# Acetaminophen

## OVERVIEW

### Introduction

Acetaminophen is a widely used nonprescription analgesic and antipyretic medication for mild-to-moderate pain and fever. Harmless at low doses, acetaminophen has direct hepatotoxic potential when taken as an overdose and can cause acute liver injury and death from acute liver failure. Even in therapeutic doses, acetaminophen can cause transient serum aminotransferase elevations.

### Background

Acetaminophen (a seet" a min' oh fen), which is known as paracetamol in Europe, is an aminophenol that is believed to act centrally as an analgesic and antipyretic agent. While technically a nonsteroidal antiinflammatory drug (NSAID), acetaminophen unlike typical NSAIDs (ibuprofen, naproxen, indomethacin) has only minor effects on tissue cyclooxygenase activity (Cox-1 and Cox-2) and appears to produce analgesia by increasing pain thresholds, perhaps through inhibition of the nitric oxide pathway which is activated by many pain neurotransmitter receptors. Acetaminophen has lower antiinflammatory activity than aspirin or typical NSAIDs. Acetaminophen is typically recommended for management of minor aches and pains from the common cold, viral and bacterial infections, sinusitis, headache, toothache, back ache, muscle strain, tendonitis, osteoarthritis, trauma or menstrual cramps. Acetaminophen has been available as an over-the-counter preparation in the United States since 1960. In 2011, an intravenous formulation of acetaminophen was approved in the United States for adults and children above the age of 2 years. The recommended oral dose is 660 to 1000 mg every 4 to 6 hours, but should not to exceed 3 grams per day. Multiple generic formulations of acetaminophen are available (e.g., Tylenol, Anacin Aspirin Free, Feverall, Neopap, Panadol and Tempra) in capsules or tablets of 330 or 500 mg each. Liquid formulations for children are available in concentrations that vary from 15 to 100 mg/mL; the dosage in children should be carefully chosen and kept to less than 75 mg/kg/day. In addition, acetaminophen is a frequent component in many over-the-counter and prescription combinations with decongestants and/or antihistamines for cold and allergy symptoms, or as a sleeping aid and with other analgesics (such as oxycodone, hydrocodone, dilaudid and codeine) for moderate-to-severe forms of pain. Common products in the United States include: Tylenol-PM, Nyquil, Darvocet, Vicodin, and many others. Acetaminophen is one of the most commonly used medications in the United States and more than 25 billion doses are sold yearly.

### Hepatotoxicity

Chronic therapy with acetaminophen in doses of 4 grams daily has been found to lead to transient elevations in serum aminotransferase levels in a proportion of subjects, generally starting after 3 to 7 days, and with peak values rising above 3-fold elevated in 39% of persons. These elevations are generally asymptomatic and resolve rapidly with stopping therapy or reducing the dosage, and in some instances resolve even with continuation at full dose (Case 1).

While acetaminophen has few side effects when used in therapeutic doses, recent reports suggest that its standard use can result in severe hypersensitivity reactions including Stevens Johnson syndrome (SJS) and toxic epidermal necrolysis (TEN). Both of these syndromes can be life-threatening and both may be accompanied by evidence of liver injury. However, the hepatic involvement is usually mild and marked only by asymptomatic mild-to-moderate elevations in serum aminotransferase levels.

The best known form of hepatoxicity from acetaminophen is an acute, serious hepatocellular injury as a result of intentional or unintentional overdose. The injury is due to a direct, toxic effect of the high doses of acetaminophen. Acetaminophen hepatotoxicity most commonly arises after a suicide attempt using more than 7.5 grams (generally more than 15 grams) as a single overdose (Case 2). Hepatic injury generally starts 24 to 72 hours after the ingestion with marked elevations in serum ALT and AST (often to above 2000 U/L), followed at 48 to 96 hours by clinical symptoms: jaundice, confusion, hepatic failure and in some instances death. Evidence of renal insufficiency is also common. Serum aminotransferase levels fall promptly and recovery is rapid if the injury is not too severe. Similar injury can occur with high therapeutic or supratherapeutic doses of acetaminophen given over several days for treatment of pain and not as a purposeful suicidal overdose (Case 3). This form of acetaminophen hepatotoxicity is referred to as accidental or unintentional overdose, and usually occurs in patients who have been fasting, or are critically ill with a concurrent illness, alcoholism or malnutrition, or have preexisting chronic liver disease. Some cases of unintentional overdose occur in patients taking acetaminophen in combinations with controlled substances (oxycodone, codeine), who take more than recommended amounts over several days in attempts to control pain or withdrawal symptoms. Instances of unintentional overdose in children are often due to errors in calculating the correct dosage or use of adult sized tablets instead of child or infant formulations. Because acetaminophen is present in many products, both by prescription and over-the-counter, another problem occurs when a patient ingests full or high doses of several products unaware that several contain acetaminophen.

Likelihood score: A[HD] (well established cause of liver injury, but severe cases occur only with high doses).

### Mechanism of Injury

The mechanism of acetaminophen hepatotoxicity has been extensively analyzed in humans and in animal models. Acetaminophen is largely converted to nontoxic glucuronate or sulfate conjugates and secreted in the urine. A minor amount of acetaminophen is metabolized via the cytochrome P450 system to intermediates that can be toxic, particularly N-acetyl-p-benzoquinoneimine. Ordinarily, this intermediate is rapidly conjugated to reduced glutathione, detoxified and secreted. If levels of glutathione are low or the pathway is overwhelmed by high doses of acetaminophen, the reactive intermediate accumulates and binds to intracellular macromolecules that can lead to cell injury, usually through apoptotic pathways. Factors that increase the metabolism of acetaminophen through the P450 system (certain drugs, chronic alcohol use) or that decrease the availability of glutathione (fasting, malnutrition, alcoholism) can predispose to acetaminophen toxicity. Factors that affect downstream toxicity of acetaminophen metabolic intermediates may also affect toxicity. These factors are important in designing therapies for acetaminophen hepatotoxicity.

### Outcome and Management

The minor aminotransferase elevations that occur during chronic therapy with acetaminophen are rarely symptomatic, generally go undetected, resolve rapidly with discontinuation of acetaminophen and sometimes even with continuation at the same dose. Such transient aminotransferase elevations do not appear to have lasting effects on the liver but can cause diagnostic confusion and lead to expensive or invasive interventions. Acetaminophen overdose, in contrast, can cause a serious acute liver injury and hepatic failure that can result in death or need for emergency liver transplantation. Currently, acetaminophen is the major cause of acute liver failure in the United States, Europe and Australia. The liver injury from acetaminophen can be prevented or ameliorated by repletion of glutathione levels which can be accomplished with n-acetylcysteine (NAC), which is available in oral and intravenous forms and should be administered immediately upon diagnosis of acetaminophen overdose. A nomogram (Rumack-Matthew Nomogram) to calculate the likelihood of liver injury from acetaminophen is available that plots acetaminophen plasma concentrations against the number of hours post-ingestion that the sample was taken. Patients with plasma levels above the “treatment line” should receive either oral or intravenous NAC. Details of administration and assistance can be obtained from the U.S. National Poison Center: 1-800-222-1222. Patients who recover spontaneously from acetaminophen hepatotoxicity generally return to normal health without evidence of chronic liver injury. The nomogram is less accurate in assessing risk with chronic or unintentional overdose. Recently, tests for acetaminophen adducts have been developed that accurately reflect hepatic damage from acetaminophen overdose and are detectable after plasma acetaminophen levels fall into undetectable range. Thus, the presence of acetaminophen adducts supports the diagnosis and their absence is a reliable in excluding acetaminophen as a cause of acute liver injury (if ALT levels are still elevated).

Drug Class: Nonsteroidal Antiinflammatory Drugs

## CASE REPORTS

### Case 1. Transient serum aminotransferase elevations due to pharmacologic doses of acetaminophen.

[Modified from: Watkins PB, Kaplowitz N, Slattery JT, Colonese CR, Colucci SV, Stewart PW, Harris SC. Aminotransferase elevations in healthy adults receiving 4 grams of acetaminophen daily: a randomized controlled trial. JAMA 2006; 296: 87-93. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/16820551)]

A healthy volunteer was started on acetaminophen in a dose of 4 grams daily as a part of a randomized controlled study of the pharmacokinetics and safety of acetaminophen combinations. After 4 days, serum ALT levels began to rise and acetaminophen was stopped on day 7 when ALT levels rose above 3-fold elevated (Table). ALT levels continued to rise, peaking at a level of 575 U/L on day 11 and slowly decreasing thereafter. The patient had no history of liver disease, tested negative for hepatitis virus markers and remained asymptomatic.

#### Key Points

Medication: | Acetaminophen (4 g daily)
Pattern: | Hepatocellular (R=14) [alkaline phosphatase levels normal]
Severity: | Mild (ALT elevations without jaundice)
Latency: | 7 days
Recovery: | ~2 weeks
Other medications: | None

#### Laboratory Values

Days After Starting | Days After Stopping | ALT (U/L) | Acetaminophen Levels (mg/dL) | Other
0
1 | | 35 | 0
2 | | 35 | 4.0
3 | | 35 | 4.5
4 | | 45 | 4.0
5 | | 70 | 3.5
6 | | 80
7 | 0 | 135 | 3.0 | Acetaminophen stopped
8 | 1 | 310
9 | 2 | 470 | 0
10 | 3 | 490
11 | 4 | 575 | 0
12 | 5 | 520
13 | 6 | 420 | 0
14 | 7 | 330
15 | 8 | 260
17 | 9 | 160
18 | 10 | 130
19 | 11 | 105
Normal Values | | <40 | 0

*Estimated from Figure 3.

#### Comment

In this carefully designed and monitored, prospective, randomized controlled trial of acetaminophen therapy, 81 of 106 patients (76%) receiving acetaminophen in doses of 4 grams daily by mouth developed at least one elevation in ALT above the upper limit of normal (ULN) (i.e., >40 U/L); in 53% ALT levels peaked at greater than 2 times ULN (>80 U/L), 39% greater than 3 times (>120 U/L), 25% greater than 5 times (>200 U/L), and 8% greater than 8 times (>320 U/L). The case shown above had one of the highest elevations observed in the study. Typically, ALT levels began to rise after 3 to 7 days and remained elevated for 1 to 11 days. No patient became jaundiced and there were no clear symptoms associated with the elevations. Patients with ALT levels rising above 3 times ULN had acetaminophen stopped, but enzyme levels continued to rise for a few days as in this patient, whose ALT level was 575 U/L 5 days after stopping drug, and at a point that acetaminophen levels were undetectable. Thus, asymptomatic ALT elevations may be caused by high therapeutic doses of acetaminophen even when plasma levels are undetectable. Partially in response to this study, recommendations were made that acetaminophen be limited to no more than 3 grams daily.

### Case 2. Severe acute acetaminophen hepatotoxicity after an intentional overdose.

[Acute Liver Failure Study Group Patient #2281]

A 27 year old woman took an overdose of acetaminophen (30 tablets of 325 mg each) in a suicide attempt because of a failed relationship. The following day she was nauseated and vomited several times, but she waited another day before presenting to an emergency room, approximately 48 hours after the ingestion. She had no other significant medical problems, and denied a history of liver disease, alcohol abuse or risk factors for viral hepatitis. On presentation, she was oriented but drowsy. Her vital signs included pulse of 125/min, BP 100/65, respirations 25/min and temperature 37 ^o^C. She was mildly jaundiced, but had no rash or signs of chronic liver disease. The total serum bilirubin level was 4.4 mg/dL, ALT 3,570 U/L, AST 7,377 U/L, and alkaline phosphatase 109 U/L (Table). A urine toxicology screen was positive for benzodiazepines and cocaine. Serum acetaminophen levels were 31 mcg/mL, and serum acetaminophen adducts were positive (23.8 nmol/mL). She was admitted to the intensive care unit and given intravenous N-acetylcysteine. Tests for hepatitis A, B and C were negative as were autoantibodies. Abdominal ultrasound showed no evidence of biliary obstruction. Over the next few days, she had mild hepatic encephalopathy. She was placed on a liver transplantation waiting list, but began to improve spontaneously, and was transferred to a psychiatric service after a week in the hospital. When finally discharged several weeks later, all liver tests had returned to normal.

#### Key Points

Medication: | Acetaminophen (~10 g as a single overdose)
Pattern: | Hepatocellular (R=~100)
Severity: | Severe (jaundice, encephalopathy and INR prolongation)
Latency: | 2 days
Recovery: | ~2 weeks
Other medications: | Possibly cocaine and benzodiazepines

#### Laboratory Values

Days After Ingestion | ALT (U/L) | Bilirubin (mg/dL) | INR | Other
2 | 3570 | 4.4 | 6.9 | Admission
3 | 7372 | 4.2 | 6.6 | Encephalopathy
4 | 5139 | 4.7 | 4.0
5 | 2852 | 5.6 | 3.7
6 | 1764 | 6.3 | 3.0
7 | 1478 | 8.0 | 3.2
8 | 828 | 9.9 | 2.1 | Transferred
Normal | <42 | <1.2 | <1.2

#### Comment

Acetaminophen hepatotoxicity typically presents within 2 to 5 days of an intentional overdose, with a pattern of acute hepatocellular necrosis with striking elevations of aminotransferase levels (often above 2000 U/L and higher than typically seen with acute viral hepatitis) and signs of hepatic failure (INR elevations) despite minimal or no jaundice. Lactic dehydrogenase values are also markedly elevated. Jaundice typically worsens over the first few days, while signs of hepatic failure may improve (encephalopathy and coagulopathy). Patients may also have renal insufficiency. Late presentation (>48 hours) after a suicidal overdose is associated with severe toxicity, while early presentation (<12 to 24 hours) is associated with milder degrees or no liver injury provided the antidote, N-acetylcysteine, is given promptly on arrival.

### Case 3. Severe acetaminophen hepatotoxicity after unintentional overdose.

[Acute Liver Failure Study Group Patient #2748]

A 69 year old woman with chronic headaches taking high doses of acetaminophen and other analgesics and over-the-counter products developed drowsiness, poor appetite, nausea, vomiting and mild diarrhea. She was brought to the emergency room by her daughter who found her mother to be confused and not her usual highly functioning self. She had a history of mitral regurgitation and was taking warfarin chronically. She had no history of liver disease, alcohol use or risk factors for viral hepatitis. Medications being taken included Tylenol, Tylenol Sinus, Vicodin, and tramadol, but the amounts being taken were not clear. The patient and her daughter denied that she was suicidal. On admission, serum acetaminophen levels were 133 mg/dL. On examination, she was confused and had asterixis. Vital signs included pulse of 136/min, respirations 18/min, BP 127/64 and temperature 36.5 ^o^C. She had no signs of chronic liver disease. Serum bilirubin was 4.8 mg/dL, ALT 5,945 U/L, AST 12,476 U/L and alkaline phosphatase was normal (Table). Tests for hepatitis A and B were negative as were autoantibodies. She had antibody to hepatitis C; HCV RNA testing was not performed. Abdominal ultrasound showed no evidence of biliary obstruction. She was given intravenous N-acetylcysteine and vitamin K. Within 2 days she began to improve clinically, and she was discharged after 7 days. In follow up 2 weeks later, all liver tests were normal and warfarin was restarted.

#### Key Points

Medication: | Acetaminophen (uncertain doses)
Pattern: | Hepatocellular (R>100) [alkaline phosphatase levels normal]
Severity: | Severe (jaundice, hospitalization and signs of hepatic failure)
Latency: | 5-7 days
Recovery: | ~2 weeks
Other medications: | Warfarin, tramadol, and oxycodone

#### Laboratory Values

Days After Stopping | ALT (U/L) | Bilirubin (mg/dL) | INR | Other
0 | 5945 | 4.8 | 3.7 | Asterixis
1 | 4675 | 7.0 | 4.7
2 | 3744 | 8.4 | 3.7
3 | 1688 | 10.1 | 3.1 | Improved mentation
4 | 1365 | 11.1 | 2.9
5 | 855 | 12.1 | 2.6
6 | 630 | 12.2 | 2.0 | Discharged
Normal | <42 | <1.2 | <1.2

#### Comment

An example of unintentional or accidental acetaminophen overdose or “therapeutic misadventure” in an elderly lady who was taking several forms of acetaminophen over several days. Contributing factors may have been chronic hepatitis C, but the pattern of serum enzyme elevations and clinical course were typical of acetaminophen overdose and not likely to be due to acute viral hepatitis. While intentional overdoses are associated with ingestion of at least 10 grams of acetaminophen at one time, unintentional overdoses are usually found with ingestion of somewhat lower amounts over a 3 to 5 day period, particularly in patients with malnutrition, alcoholism, chronic liver disease or an accompanying medical illness. Cases are frequently associated with use of narcotic combinations (such as hydrocodone with acetaminophen), with abuse of the narcotic leading to increasing acetaminophen exposure. Finally, in many situations such as this case, the actual amount of acetaminophen ingested is unclear.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Acetaminophen – Generic, Various Trade Names

DRUG CLASS

Nonsteroidal Antiinflammatory Drugs

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Acetaminophen)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Acetaminophen | 103-90-2 | C8-H9-N-O2 | Acetaminophen Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 28 January 2016

Zimmerman HJ. Acetaminophen (Paracetamol). In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 271-4 and 540-1. (Expert review of acetaminophen hepatotoxicity published in 1999).
Hinson JA. Mechanisms of acetaminophen-induced liver disease. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 305-30. (Review of the mechanisms of liver cell injury due to acetaminophen published in 2007).
James LP. Acetaminophen. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 331-42. (Review of the clinical and pathological features and diagnosis of acetaminophen-hepatotoxicity).
Grosser T, Smyth E, FitzGerald GA. Para-Aminophenol derivatives: acetaminophen. Anti-inflammatory, antipyretic and analgesic agents; pharmacology of gout. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 982-4. (Textbook of pharmacology and therapeutics).
Davidson DG, Eastham WN. Acute liver necrosis following overdose of paracetamol. Br Med J 1966; 2: 497-9. (Two cases of fatal acute liver failure with hypoglycemia after acetaminophen overdose [17 and 50 g]; marked centrilobular hepatic necrosis found histologically: early report). 5913083
Thompson JS, Prescott LF. Br Med J 1966; 2: 506-7. (54 year old man took an overdose of ~23 g of acetaminophen and developed drowsiness followed by jaundice 6 days later [bilirubin 4.4 mg/dL, ALT 124 U/L], recovering spontaneously: early report). 5913085
Clark R, Borirakchanyavat V, Davidson AR, Thompson RP, Widdop B, Goulding R, Williams R. Hepatic damage and death from overdose of paracetamol. Lancet 1973; 1: 66-70. (Among 60 patients with acetaminophen overdose, 49 developed liver damage, 17 hepatic failure, and 12 died. Biopsies showed centrilobular necrosis and collapse; prognosis correlated with protime and bilirubin levels; increasing number of cases were found between 1966 and 1971). 4118649
Mitchell JR, Thorgeirsson SS, Potter WZ, Jollow DJ, Keiser H. Acetaminophen-induced hepatic injury: protective role of glutathione in man and rationale for therapy. Clin Pharmacol Ther 1974; 16: 676-84. (Analysis of metabolites of acetaminophen in humans and mice; mercapturic acid ordinarily detoxified by conjugation to glutathione; study demonstrating basis for use of glutathione-like nucleophiles for acetaminophen toxicity). 4417718
McJunkin B, Barwick KW, Little WC, Winfield JB. Fatal massive hepatic necrosis following acetaminophen overdose. JAMA 1976; 236: 1874-5. (24 year old woman took overdose of 13 g of acetaminophen and developed acute liver failure and death in 7 days [bilirubin 11.9 mg/dL, AST 8795 U/L, Alk P 189 U/L, LDH >2400 U/L, protime 72 sec]; early report from US). 989539
Ambre J, Alexander M. Liver toxicity after acetaminophen ingestion. Inadequacy of the dose estimate as an index of risk. JAMA 1977; 238: 500-1. (Clinical history of amount of acetaminophen ingested may be inaccurate; 5 cases in which a significant overdose was reported by the patient with only low levels of acetaminophen found in plasma and no subsequent liver injury). 577576
Rumack BH, Peterson RG. Acetaminophen overdose: incidence, diagnosis, and management in 416 patients. Pediatrics 1978; 62(5 Pt 2 Suppl): 898-903. (Nationwide multicenter study identified 25% of acetaminophen overdoses [112/416] as having "toxic" levels; no deaths among 100 patients treated with N-acetylcysteine within 24 hours of ingestion). 724342
Licht H, Seeff LB, Zimmerman HJ. Apparent potentiation of acetaminophen hepatotoxicity by alcohol. Ann Intern Med 1980; 92: 511-6. (53 year old alcoholic man with chronic intermittent use of 2.5-3.9 g of acetaminophen daily developed acute liver injury and ascites [bilirubin 13 mg/dL, ALT 4560 U/L, protime 22 sec], recovering spontaneously). 7362155
Rumack BH, Peterson RG, Koch GG, Amara IA. Acetaminophen overdose: 662 cases with evaluation of oral acetylcysteine treatment. Arch Intern Med 1981; 141: 380-5. (Among 662 patients with acetaminophen overdose in a national open-clinic study, no deaths occurred if N-acetylcysteine [NAC] was given within 24 hours; among those with toxic levels, AST elevations above 1000 U/L occurred in 7% given NAC within 10 hours, 29% at 10-16 hours, and 62% at 16-24 hours). 7469629
Black M, Cornell JF, Rabin L, Shachter N. Late presentation of acetaminophen hepatotoxicity. Dig Dis Sci 1982; 27: 370-4. (37 year old woman with chronic alcoholism took 10 g acetaminophen daily for several weeks and developed acute liver failure [bilirubin 3.9 rising to 19 mg/dL, AST 13,350 U/L] and death; recognition of role of acetaminophen was delayed; autopsy showed centrilobular necrosis and steatohepatitis). 7067588
Byer AJ, Traylor TR, Semmer JR. Acetaminophen overdose in the third trimester of pregnancy. JAMA 1982; 247: 3114-5. (26 year old woman took overdose of acetaminophen [22.5 g] at 36 weeks gestation and was given N-acetylcysteine within <10 hours and had no subsequent ALT elevations; uneventful delivery and normal child 6 weeks later). 7077806
Benson GD. Acetaminophen in chronic liver disease. Clin Pharmacol Ther 1983; 33: 95-101. (Six patients with chronic liver disease were given 4.0 g/day of acetaminophen for 5 days without evidence of drug accumulation or ALT elevations; 20 patients given 4 g acetaminophen or placebo for 13 days, with no differences in two groups). 6848304
Haibach H, Akhter JE, Muscato MS, Cary PL, Hoffmann MF. Acetaminophen overdose with fetal demise. Am J Clin Pathhol 1984; 82: 240-2. (24 year old woman presented 15-39 hours after overdose of acetaminophen at 28 week gestation [bilirubin not given, ALT 1410 rising to 4521 U/L], and dead fetus, autopsy of infant showing massive "cytolysis"). 6465090
Rumack BH. Acetaminophen overdose in young children: treatment and effects of alcohol and other additional ingestants in 417 cases. Am J Dis Child 1984; 138: 428-33. (417 children with acetaminophen overdose in multicenter study; 55 with a toxic level; 43 treated with N-acetylcysteine; no deaths; those with other ingestants had more lethargy and higher AST levels). 6711498
Seeff LB, Cuccherini BA, Zimmerman HJ, Adler E, Benjamin SB. Acetaminophen hepatotoxicity in alcoholics. A therapeutic misadventure. Ann Intern Med 1986; 104: 399-404. (6 case reports and review of 19 cases in literature on acetaminophen toxicity in alcoholics taking 2.6-16.5 g daily for pain or fever [bilirubin 1.3-35 mg/dL, AST 2870-26,900 U/L], all survived). 3511825
Smilkstein MJ, Knapp GL, Kulig KW, Rumack BH. Efficacy of oral N-acetylcysteine in the treatment of acetaminophen overdose: analysis of the National Multicenter Study(1976-1985). N Engl J Med 1988; 319: 1557-62. (Results of multicenter trial of 2540 patients with acetaminophen overdose given NAC: 28 deaths due to acetaminophen, but none among those given N-acetylcysteine [NAC] less than 16 hours after overdose; rate of ALT >1000 U/L was 6% if NAC given within 10 hours, 26% if between 10 and 24 hours after ingestion). 3059186
Foust RT, Reddy KR, Jeffers LJ, Schiff ER. Nyquil-associated liver injury. Am J Gastroenterol 1989; 84: 422-5. (56 year old man and 37 year old woman developed acute liver failure after ingestion of bottle of Nyquil [420 mL: 14 g acetaminophen in 25% alcohol] over 1-3 days [bilirubin 1.3 and 12.5 mg/dL, AST 8285 and 2413 U/L, Alk P 249 and 53 U/L], both survived). 2929565
Harrison PM, Keays R, Bray GP, Alexander GJM, Williams R. Improved outcome of paracetamol-induced fulminant hepatic failure by late administration of acetylcysteine. Lancet 1990; 335: 1572-3. (Retrospective analysis of 100 patients with acetaminophen induced acute liver failure found lower mortality in those receiving N-acetylcysteine [NAC] 10-36 hours after overdose than controls [37% vs 58%], suggesting beneficial effects of NAC even if given somewhat late). 1072496
Wootton FT, Lee WM. Acetaminophen hepatotoxicity in the alcoholic. South Med J 1990; 83: 1047-9. (In retrospective review from a single center over 2 years, 7 cases of suspected acetaminophen hepatotoxicity were identified among alcoholics taking high or super-therapeutic doses [3.5-11 g daily for 2-6 days], all with high AST [4472-21660 U/L] and 3 fatal). 2402650
Keays R, Harrison PM, Wendon JA, Forbes A, Gove C, Alexander GJM, Williams R. Intravenous acetylcysteine in paracetamol induced fulminant hepatic failure: a prospective controlled trial. BMJ 1991; 303: 1026-9. (Randomized controlled trial of intravenous N-acetylcysteine [NAC] vs no therapy in 50 patients with acute liver failure 36 to 80 hours after acetaminophen overdose found improved survival [48% vs 20%] and less cerebral edema, suggesting that late administration of NAC is partially effective). 1954453
Whitcomb DC, Block GD. Association of acetaminophen hepatotoxicity with fasting and ethanol use. JAMA 1994; 272: 1845-50. (Retrospective analysis of 49 patients presenting with acetaminophen hepatotoxicity at single center over 7 years; 43% of cases were unintentional with doses of 4-10 g daily, often in context of recent fasting rather than alcoholism). 7990219
Cassidy WM, Reynolds TB. Serum lactic dehydrogenase in the differential diagnosis of acute hepatocellular injury. J Clin Gastroenterol 1994; 19: 118-21. (Retrospective review of 97 cases of acute liver injury for lactic dehydrogenase [LDH] levels; marked and similar elevations of LDH and ALT or AST found in ischemic hepatitis and acetaminophen toxicity compared to viral hepatitis). 7963356
Bonkovsky HL, Kane RE, Jones DP, Galinsky RE, Banner B. Acute hepatic and renal toxicity from low doses of acetaminophen in the absence of alcohol abuse or malnutrition: evidence for increased susceptibility to drug toxicity due to cardiopulmonary and renal insufficiency. Hepatology 1994; 19: 1141-8. (67 year old man with severe pulmonary and cardiovascular disease developed acute liver injury after taking 1-3 g of acetaminophen daily for 2 days [bilirubin 2.7 mg/dL, ALT 2175 U/L, LDH 3125 U/L, Alk P 130 U/L], resolving rapidly; role of acute ischemic hepatitis could not be excluded). 8175135
Makin AJ, Wendon J, Williams R. A 7-year experience of severe acetaminophen-induce hepatotoxicity(1987-1993). Gastroenterology 1995; 109: 1907-16. (7 year experience from King's College Hospital acute liver failure group of 560 patients with acetaminophen hepatotoxicity, rate increased over time [58 to 123 cases yearly], but survival improved [<50% to 78%] while use of N-acetylcysteine [NAC] [40% to 83%] and transplant [1 to 13 per year] increased; 8% were considered accidental or unintentional). 7820317
Alonso EM, Sokol RJ, Hart J, Tyson RW, Narkewicz MR, Whitington PF. Fulminant hepatitis associated with centrilobular hepatic necrosis in young children. J Pediatr 1995; 127: 888-94. (7 children with prodrome of viral illness followed by encephalopathy, liver injury, mild jaundice and centrilobular necrosis; cause was not identified, but authors thought that course was worsened by acetaminophen). 8523184
Zimmerman HJ, Maddrey WC. Acetaminophen(paracetamol) hepatotoxicity with regular intake of alcohol: analysis of instances of therapeutic misadventure. Hepatology 1995; 22: 767-73. (Analysis of 67 patients enrolled in registry of alcoholic patients with unintentional acetaminophen toxicity usually taking it for pain or fever, in doses of <4 to >15 g daily for 1 to 30 days; 18% fatal; AST >3000 U/L in 90%; similar features in 94 cases in literature). 7657281
Schiodt FV, Rochling FA, Casey DL, Lee WM. Acetaminophen toxicity in an urban county hospital. N Engl J Med 1997; 337: 1112-7. (Retrospective analysis of 71 patients admitted to Parkland Memorial Hospital, Dallas for acetaminophen overdose between 1992-5 found 50 due to single suicidal dose and 21 due to unintentional overdose, typically while attempting to control pain. Accidental cases were more severe, older, more likely alcoholic, more often using other analgesics and had higher mortality rate [19% vs 2%]). 9329933
Johnston SC, Pelleier LL, Jr. Enhanced hepatotoxicity of acetaminophen in the alcoholic patient: two case reports and a review of the literature. Medicine (Baltimore) 1997; 76: 185-91. (43 year old male and 46 year old female alcoholic taking 7.1 and 7.7 g acetaminophen over 24 hours for pain developed acute liver failure and died [bilirubin 13 mg/dL and not given, AST 8,685 and 14,000 U/L, protime 32.8 and 44.2 sec]; literature review of 51 cases of unintentional acetaminophen overdose in alcoholics). 9193453
Thomas SH, Horner JE, Chew K, Connolly J, Dorani B, Bevan L, Bhattacharyya S, et al. Paracetamol poisoning in the north east of England: presentation, early management and outcome. Hum Exp Toxicol 1997; 16: 495-500. (Among 400 presentations of acute acetaminophen overdose, serum levels at 4 hours correlated only weakly with reported dose and were above the normogram treatment line in 20% of those who reported taking more than 12 g and in 3% of those taking less). 9306135
Andrade RJ, Lucena MI, Garcia-Escano D, Camargo R. Severe idiosyncratic acute hepatic injury caused by paracetamol. J Hepatol 1998; 28: 1078. (29 year old woman developed jaundice [bilirubin 13.9 mg/dL, ALT 945 U/L, Alk P 532 U/L] 11 days after 7 day course of roxithromycin and acetaminophen [1.5 g daily], recovering in 2 months; restarting acetaminophen [~1 g/day for 2 days] was followed by acute rise in ALT to 3216 U/L but normal bilirubin, resolving rapidly; interpreted initial episode as due to roxithromycin, with increased susceptibility to acetaminophen during recovery). 9672188
Gow PJ, Smallwood RA, Angus PW. Paracetamol overdose in a liver transplantation centre: an 8-year experience. J Gastroenterol Hepatol 1999; 14: 817-21. (Retrospective review of 152 patients with acetaminophen overdose from an Australian center found increasing rate in population, 29 patients had hepatotoxicity, 13 developed acute liver failure, one had liver transplant and subsequently died, no other fatalities). 10482436
Bond GR, Hite LK. Population-based incidence and outcome of acetaminophen poisoning by type of ingestion. Acad Emerg Med 1999; 6: 115-20. (Retrospective analysis of patients admitted to four hospitals over 4 years; 137 cases of acetaminophen overdose, 5.5 per 100,000 person-years, rarely serious and often too late for use of nomogram). 10569383
Alander SW, Dowd MD, Bratton SL, Kearns GL. Pediatric acetaminophen overdose: risk factors associated with hepatocellular injury. Arch Pediatr Adolesc Med 2000; 154: 346-50. (Retrospective analysis of 322 children with acetaminophen overdose from two centers between 1988 and 1997; ALT elevations in 8%, liver failure in 4 [1%], and 1 death; overdose was unintentional in 54% [ages 2 months to 13 years], only one case of which led to liver injury [0.6%] and none to liver failure). 10768670
Broughan TA, Soloway RD. Acetaminophen hepatoxicity. Dig Dis Sci 2000; 45: 1553-8. (Retrospective chart review found 48 cases of acetaminophen hepatotoxicity admitted to single hospital over 7 year period: 8 unintentional; 2 fatalities, 1 transplanted). 11007105
Caravati EM. Unintentional acetaminophen ingestion in children and the potential for hepatotoxicity. Clin Toxicol 2000; 38: 291-6. (Prospective evaluation of 1015 children with single acetaminophen overdose of >140 mg/kg; only 8 [ages 1-2 years] had potentially hepatotoxic plasma levels, all had received >200 mg/kg [5 received adult formulation], suggesting that lower ingestions can be treated at home). 10866329
Cranswick N, Coghlan D. Paracetamol efficacy and safety in children: the first 40 years. Am J Ther 2000; 7: 135-41. (Review of use, efficacy and safety of acetaminophen in children). 11319581
Ostapowicz G, Lee WM. Acute hepatic failure: a Western perspective. J Gastroenterol Hepatol 2000; 15: 480-8. (Review of acute liver failure contrasting experience in different areas of the world, more diverse causes in the West including drug induced liver disease in 7-16%, acetaminophen 58% in the UK and 20% in US, but <2% in France, Australia and India). 10847432
Halevi A, Ben-Amitai D, Garty BZ. Toxic epidermal necrolysis associated with acetaminophen ingestion. Ann Pharmacother 2000; 34: 32-4. (7 year old girl developed toxic epidermal necrolysis [TEN] 12 hours after receiving 3 doses of acetaminophen for fever and sore throat [eosinophils 8%, bilirubin not given, ALT 88 U/L, AST 55 U/L, CK 1660 U/L], later developing erythema, urticaria, fever and hypotension 30 minutes after a single challenge dose). 10669183
Makin A, Williams R. Paracetamol hepatotoxicity and alcohol consumption in deliberate and accidental overdose. Q J Med 2000; 93: 314-9. (Retrospective analysis of 553 case of acetaminophen hepatoxicity seen at King's College Hospital over 7 years, 38 [7%] were unintentional, alcohol use more common with accidental overdose but heavy use more common in suicidal group; no correlation of alcohol with severity). 10873183
Kuffner EK, Dart RC, Bogdan GM, Hill RE, Casper E, Darton L. Effect of maximal daily doses of acetaminophen on the liver of alcoholic patients: a randomized, double-blind, placebo-controlled trial. Arch Intern Med 2001; 161: 2247-52. (201 patients enrolled in randomized controlled trial of 4 g of acetaminophen for 2 days in patients entering alcohol rehabilitation program found no significant changes in ALT or AST levels, minor elevations were similar in frequency in both groups). 11575982
Bareille MP, Montastruc JL, Lapeyre-Mestre M. [Liver damage and nonsteroidal anti-inflammatory drugs: case non-case study in the French Pharmacovigilance Database] Therapie 2001; 56: 51-5. French. (Comparing adverse event reports designated as liver related or not found increased rate of liver related reports attributed to acetaminophen). 11322018
Caravati EM. Safety of childhood acetaminophen overdose. Ann Emerg Med 2001; 37: 114-6. (Letter raising the issue of minimum acute hepatotoxic dose of acetaminophen in children suggesting that 200 mg/kg may be too high). 11145785
Farooqi VA, Khokhar N. Paracetamol poisoning resulting in massively raised serum transaminases. J Pak Med Assoc 2001; 51: 303-4. (45 year old British woman took 15 g overdose of acetaminophen while visiting in Pakistan and presented with ALT values of 1121 U/L, rising to 14,544 2 days later; given N-acetylcysteine and recovered). 11715899
Ganry H, Pruvot F, Vesque D, Schmidely N. [Liver and renal tolerance to paracetamol: 3 g or 4 g per day?]. Presse Med 2001; 30: 724-30. French. 1136073
James LP, Wilson JT, Simar R, Farrar HC, Kearns GL, Simposon PM, Hinson JA, et al., Pediatric Pharmacology Research Unit Network. Evaluation of occult acetaminophen hepatotoxicity in hospitalized children receiving acetaminophen. Clin Pediatr(Phila) 2001; 40: 243-8. (Acetaminophen adducts were highly specific for acetaminophen induced hepatic injury in animal models; immunoblot assay for adducts however, identified them in only 1 of 12 children with hepatotoxicity after overdose). 11388672
Shinzawa H, Togashi H, Sugahara K, Ishibashi M, Terui Y, Aoki M, Mitsuhashi H, et al. Acute cholestatic hepatitis caused by a probable allergic reaction to paracetamol in an adolescent. Tohoku J Exp Med 2001; 193: 255-8. (14 year old girl developed rash and acute liver injury after few days of acetaminophen, but also taking midecamycin [bilirubin 2.4 rising to 12.4 mg/dL, ALT 512 U/L, Alk P 1930 U/L, 12% eosinophilia], suffering prolonged jaundice which required prednisone therapy; positive lymphocyte stimulation test to acetaminophen). 11315774
Sztajnkrycer MJ, Bond GR. Chronic acetaminophen overdosing in children: risk assessment and management. Curr Opin Pediatr 2001; 13: 177-82. (Review of diagnosis and management of acetaminophen overdose in children). 11317062
Gill EJ, Contos MJ, Peng TC. Acute fatty liver of pregnancy and acetaminophen toxicity leading to liver failure and postpartum liver transplantation. A case report. J Reprod Med 2002; 47: 584-6. (18 year old woman with acute fatty liver of pregnancy at 33 weeks gestation with fetal death and hepatic failure [ALT 4112 U/L] and vague history of acetaminophen intake; liver biopsy showed both centrolobular necrosis and microvesicular fatty change; patient underwent liver transplantation). 12170538
Prandota J. Important role of prodromal viral infections responsible for inhibition of xenobiotic metabolizing enzymes in the pathomechanism of idiopathic Reye's syndrome, Stevens-Johnson syndrome, autoimmune hepatitis, and hepatotoxicity of the therapeutic doses of acetaminophen used in genetically predisposed persons. Am J Ther 2002; 9: 149-56. (Review article suggesting that viral infections may predispose to several syndromes including Reye and Stevens Johnson syndrome, autoimmune hepatitis, and acetaminophen hepatotoxicity). 11897929
Gyamlani GG, Parikh CR. Acetaminophen toxicity: suicidal vs. accidental. Crit Care 2002; 6: 155-9. (Among 93 patients with acetaminophen toxicity seen over 52 month period, 13 were accidental and levels were not as predictive of liver injury as in 80 suicidal cases; 2 deaths in accidental group). 11983042
Lukasik-Glebocka M, Klimaszyk D. [Alcohol-paracetamol syndrome: a case report] Przegl Lek 2002; 59: 381-3. Polish. 1218401
Ostapowicz G, Fontana RJ, Schiodt FV, Larson A, Davern TJ, Han SH, McCashland TM, et al.; U.S. Acute Liver Failure Study Group. Results of a prospective study of acute liver failure at 17 tertiary care centers in the United States. Ann Intern Med 2002; 137: 947-54. (Analysis of 308 cases of acute liver failure seen at 17 centers over 3.5 year period; acetaminophen was cause of 38%; in comparison to others, patients with acetaminophen injury were typically younger, more often white, had higher survival without transplant [68%], shorter time from jaundice to encephalopathy, higher mean ALT and AST levels and lower bilirubin levels). 12484709
Rumack BH. Acetaminophen hepatotoxicity: the first 35 years. J Toxicol Clin Toxicol 2002; 40: 3-20. (Personal review of development of the nomogram for acetaminophen hepatotoxicity and its therapy with N-acetylcysteine, evolution of understanding of the mechanism of liver injury, the role of CPY2E1 and issues in interpretation of acetaminophen ingestion history and plasma levels). 11990202
Schmidt LE, Dalhoff K. Serum phosphate is an early predictor of outcome in severe acetaminophen-induced hepatotoxicity. Hepatology 2002; 36: 659-65. (High phosphate levels were more common among patients with acetaminophen hepatotoxicity and among fatal than nonfatal cases, perhaps reflecting renal insufficiency). 12198658
Schiodt FV, Lee WM, Bondesen S, Ott P, Christensen E. Influence of acute and chronic alcohol intake on the clinical course and outcome in acetaminophen overdose. Aliment Pharmacol Ther 2002; 16: 707-15. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/%2011929388) (Among 209 patients admitted to Copenhagen hospital with acetaminophen overdose between 1993-6, analysis showed that chronic alcohol intake and delay to N-acetylcysteine [NAC] treatment were associated with severe course, but only delay to NAC with decreased survival).
Bolesta S, Haber SL. Hepatotoxicity associated with chronic acetaminophen administration in patients with risk factors. Ann Pharmacother 2002; 36: 331-3. (Literature review found 4 case reports of liver toxicity with acetaminophen doses of <4 g daily and no risk factors; these instances were marked mostly by AST elevations only and several had other possible causes of liver disease). 11847957
Kurtovic J, Riordan SM. Paracetamol-induced hepatotoxicity at recommended dosage. J Intern Med 2003; 253: 240-3. (53 year old woman on chemotherapy, who had malnutrition and was fasting, developed acute hepatic injury on acetaminophen 4 g daily while in hospital [bilirubin 1.8 mg/dL, ALT 5920 U/L, Alk P 169 U/L], resolving with NAC therapy; no recurrence on rechallenge with lower doses). 12542566
Fukumoto M. [Acetaminophen poisoning] Chudoku Kenkyu 2003; 16: 285-97. Japanese. 1458235
Heaton PC, Cluxton RJ Jr, Moomaw CJ. Acetaminophen overuse in the Ohio Medicaid population. J Am Pharm Assoc 2003; 43: 680-4. (Analysis of Medicaid claims data demonstrating that 3% of prescriptions were for high therapeutic doses of acetaminophen in patients with liver disease). 14717264
James LP, Mayeux PR, Hinson JA. Acetaminophen-induced hepatotoxicity. Drug Metab Dispos 2003; 31: 1499-506. (Review of metabolism of acetaminophen and mechanisms of hepatotoxicity). 14625346
Kociancic T, Reed MD. Acetaminophen intoxication and length of treatment: how long is long enough? Pharmacotherapy 2003; 23: 1052-9. (Current regimen of oral NAC is 140 mg/kg followed by 70 mg/kg every 4 hours for 17 doses [total of 72 hours]; shorter courses would be easier and less expensive). 12921251
McGregor AH, More LJ, Simpson KJ, Harrison DJ. Liver death and regeneration in paracetamol toxicity. Hum Exp Toxicol 2003; 22: 221-7. (Histology of acetaminophen hepatotoxicity reveals apoptosis in 0.6% of cells, suggesting role of programmed cell death in injury). 12755473
Lee WM. Acetaminophen and the U.S. Acute Liver Failure Study Group: lowering the risks of hepatic failure. Hepatology 2004; 40: 6-9. (Editorial on burden of acetaminophen poisoning in the US, raising issue of limitation of the availability of acetaminophen as an over-the-counter agent). 15239078
Davern TJ 2nd. Acetaminophen hepatotoxicity. Hepatology 2004; 40: 1021-2; discussion 1022. 1538215
Parikh S, Dillon LC, Scharf SL. Hepatotoxicity possibly due to paracetamol with carbamazepine. Intern Med J 2004; 34: 441-2. (80 year old woman with dementia given 4 g acetaminophen daily for 18 days developed liver injury [bilirubin 0.8 rising to 3.6 mg/dL, ALT 974 U/L, Alk P 161 U/L], resolving rapidly with NAC therapy). 15271182
Bygum A, Gregersen JW, Buus SK. Acetaminophen-induced toxic epidermal necrolysis in a child. Pediatr Dermatol 2004; 21: 236-8. . (6 year old boy developed toxic epidermal necrolysis [TEN] affecting 50-60% of body surface with a prolonged complicated course; later information was provided that he had taken acetaminophen daily for the 2 weeks before onset). 15165202
Shaoul R, Novikov J, Maor I, Jaffe M. Silent acetaminophen-induced hepatotoxicity in febrile children: does this entity exist? Acta Paediatr 2004; 93: 618-22. (Prospective study of 107 children given acetaminophen during febrile illness; no correlation found between dose or plasma levels of acetaminophen with elevations in ALT or AST levels). 15174783
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug induced liver injury in the United States. Liver Transplant 2004; 10: 1018-23. (Analysis of 12 years of UNOS data found that 15% of liver transplants done for acute liver failure in the US were for drug induced liver disease, half attributed to acetaminophen, including 15 of 41 pediatric transplants). 15390328
Ayonrinde OT, Phelps GJ, Hurley JC, Ayonrinde OA. Paracetamol overdose and hepatotoxicity at a regional Australian hospital: a 4-year experience. Intern Med J 2005; 35: 655-60. (Retrospective review of 192 cases of acute acetaminophen toxicity from a single Australian hospital found rising rates of overdose; 26 [13%] with hepatotoxicity, severe in 6 [3%], concurrent alcohol use did not correlate with severity of liver injury). 16248859
Björnsson E, Jerlstad P, Bergqvist A, Olsson R. Fulminant drug-induced hepatic failure leading to death or liver transplantation in Sweden. Scand J Gastroenterol 2005; 40: 1095-101. (36 years of reporting to Swedish registry identified 103 cases of acute liver failure due to drugs; acetaminophen accounting for 14 [14%] and being the second most common cause, after halothane). 16165719
Dart RC, Green JL, Bogdan GM. The safety profile of sustained release paracetamol during therapeutic use and following overdose. Drug Saf 2005; 28: 1045-56. (Literature search and analysis of poison center database indicated that sustained release forms of acetaminophen have similar safety and toxicity profile to standard acetaminophen, although nomogram may not be as accurate and levels may rise during monitoring). 16231956
Graham GG, Scott KF, Day RO. Tolerability of paracetamol. Drug Saf 2005; 28: 227-40. (Review on tolerability of acetaminophen which concludes that "critical analysis indicates that most patients with alleged toxicity from therapeutic doses have taken overdoses"). 15733027
Wilkes JM, Clark LE, Herrera JL. Acetaminophen overdose in pregnancy. South Med J 2005; 98: 1118-22. (Review; acetaminophen can cross the placenta and cause hepatic injury in fetal liver; NAC crosses placenta as well). 16351032
Larson AM, Polson J, Fontana RJ, Davern TJ, Lalani E, Hynan LS, Reisch JS, et al., Acute Liver Failure Study Group. Acetaminophen-induced acute liver failure: results of a United States Multicenter, Prospective Study. Hepatology 2005; 42: 1364-72. (In a 6 year study at 22 US centers, 275 of 662 cases [42%] of acute liver failure were due to acetaminophen, accounting for 1/3rd of deaths; frequency increased over time from 28%-51%; 65% spontaneous survival, 8% transplanted, 27% died; about half were unintentional, with average total dose of 20 vs 25 g exposure; similar course and outcome to intentional overdose cases). 16317692
Björnsson E, Olsson R. Suspected drug-induced liver fatalities reported to the WHO database. Dig Liver Dis 2006; 38: 33-8. (In WHO database of fatal adverse drug reactions from 1968-2003, there were 4690 reports of drug induced liver fatality, acetaminophen being the most common cause [>300 cases: but 93% were reported from the US). 16054882
Kozer E, Greenberg R, Zimmerman DR, Berkovitch M. Repeated supratherapeutic doses of paracetamol in children - a literature review and suggested clinical approach. Acta Paediatr 2006; 95: 1165-71. (Review stressing the rarity of liver injury from acetaminophen in children, reported largely by hepatology referral centers, but rarely seen in cohort studies of acetaminophen overdoses; recommended using <75 mg/kg/day as a safe dose in children). 16982484
Kuffner EK, Temple AR, Cooper KM, Baggish JS, Parenti DL. Retrospective analysis of transient elevations in alanine aminotransferase during long-term treatment with acetaminophen in osteoarthritis clinical trials. Curr Med Res Opin 2006; 22: 2137-48. (Retrospective analysis of ALT results from 7 trials using acetaminophen [1950-4000 mg/day for 4-12 weeks, one for 12 months] for osteoarthritis, found no cases of hepatotoxicity or hepatic failure; 17% of participants had ALT elevation, but none >3 times ULN and high bilirubin; all resolved, some despite continuation of acetaminophen at previous dose). 17076974
James LP, Alonso EM, Hynan LS, Hinson JA, Davern TJ, Lee WM, Squires RH, Pediatric Acute Liver Failure Study Group. Detection of acetaminophen protein adducts in children with acute liver failure of indeterminate cause. Pediatrics 2006: 118: e676-e681. (N-acetylbenzquinoneimine metabolite of acetaminophen binds to cysteine residues of proteins and can be detected in serum with HPLC-EC; testing of 104 children with acute liver failure identified adducts in 90% of cases attributed to acetaminophen, but also in 9% of cases of other known cause and 12.5% of indeterminate cause; these cases having clinical features resembling acetaminophen hepatic injury). 16950959
Davern TJ 2nd, James LP, Hinson JA, Polson J, Larson AM, Fontana RJ, Lalani E, et al.; Acute Liver Failure Study Group. Measurement of serum acetaminophen-protein adducts in patients with acute liver failure. Gastroenterology 2006; 130: 687-94. (Acetaminophen-protein adducts detected in all 20 cases of acetaminophen induced acute liver failure in adults, but also in 19% [7/36] of cases of indeterminate cause; adduct levels fell in parallel with ALT, and long after acetaminophen was no longer detected by routine tests). 16530510
Mahadevan SB, McKiernan PJ, Davies P, Kelly DA. Paracetamol induced hepatotoxicity. Arch Dis Child 2006; 91: 598-603. (Analysis of 51 children with acetaminophen hepatotoxicity admitted to a single center from 1992-2002, 45 with single overdose, 6 with chronic use [<7 years]; 21 developed acute liver failure with encephalopathy; all with grade III encephalopathy either died [n=5] or underwent liver transplant [n=6]). 16547087
Moling O, Cairon E, Rimenti G, Rizza F, Pristerá, Mian P. Severe hepatotoxicity after therapeutic doses of acetaminophen. Clin Ther 2006; 28: 755-60. (45 year old man with HIV, HBV and HCV co-infection developed hepatic injury after taking 4 g of acetaminophen daily for 4 days for fever [bilirubin 2.3 mg/dL, ALT 5433 U/L, LDH 13,641 U/L, INR 2.1], recovering rapidly after N-acetylcysteine). 16861097
Ranganathan SS, Sathiadas MG, Sumanasena S, Fernandopulle M, Lamabadusuriya SP, Fernandopulle BM. Fulminant hepatic failure and paracetamol overuse with therapeutic intent in febrile children. Indian J Pediatr 2006; 73: 871-5. (All 25 children with acute liver failure presenting at a hospital in Colombo, Ski Lanka compared to only 33% of 33 hospitalized controls had consumed acetaminophen before presentation). 17090896
Brok J, Buckley N, Gluud C. Interventions for paracetamol(acetaminophen) overdose. Cochrane Database Syst Rev 2006;(2): CD003328. (Systematic review of literature on interventions for acetaminophen overdose, supports use of N-acetylcysteine; activated charcoal delays absorption of acetaminophen, but its efficacy in decreasing injury is unclear). 16625578
Watkins PB, Kaplowitz N, Slattery JT, Colonese CR, Colucci SV, Stewart PW, Harris SC. Aminotransferase elevations in healthy adults receiving 4 grams of acetaminophen daily: a randomized controlled trial. JAMA. 2006; 296: 87-93. (Randomized controlled trial of acetaminophen [4 g daily for 14 days] in combination with various other analgesics versus placebo in 134 healthy controls found elevations in ALT levels to be common with acetaminophen and not affected by the combination with other agents: ALT levels rose above 3 times ULN in 39%, >5 times in 25% and >8 times in 8%; no patient had symptoms or became jaundiced, and elevations resolved rapidly with discontinuation: Case #1). 16820551
Yuan Y, Thabane M, Thabane L, Hunt RH. Acetaminophen and aminotransferase elevations. JAMA 2006; 296: 2798; author reply 2798-9. (Letter in response to Watkins et al. [2006] raising statistical and design issues without new information). 17179451
Khashab M, Tector AJ, Kwo PY. Epidemiology of acute liver failure. Curr Gastroenterol Rep 2007; 9: 66-73. (Review of frequency and major causes of acute liver failure). 17335680
Brune K, Nitschmann S. [Liver toxicity of paracetamol] Internist(Berl) 2007; 48: 1036-8. German. 1771253
Dart RC, Bailey E. Does therapeutic use of acetaminophen cause acute liver failure? Pharmacotherapy 2007; 27: 1219-30. (Analysis of literature on safety of high but therapeutic doses of acetaminophen: among 30,865 patients followed prospectively, no case of acute liver failure was identified and only 0.4% of patients had ALT levels above the ULN [often similar to rate in controls]; among 9,337 patients in retrospective studies, 1.0% had ALT elevations and 0.07% had acute liver failure, some of whom may have taken higher than prescribed doses). 17723075
Dart RC, Rumack BH. Patient-tailored acetylcysteine administration. Ann Emerg Med 2007; 50: 280-1. . (Editorial discussing difficulties of shortening the course of N-acetylcysteine therapy based upon response). 17418449
Escorsell A, Mas A, de la Mata M; Spanish Group for the Study of Acute Liver Failure. Acute liver failure in Spain: analysis of 267 cases. Liver Transpl 2007; 13: 1389-95. (In Spain, acetaminophen hepatotoxicity is uncommon, accounting for only 6 of 267 cases [2%] of acute liver failure identified at 17 referral hospitals between 1992 and 2000; other causes included HBV in 29%, other drugs in 20%). 17370334
Heard K, Green JL, Bailey JE, Bogdan GM, Dart RC. A randomized trial to determine the change in alanine aminotransferase during 10 days of paracetamol(acetaminophen) administration in subjects who consume moderate amounts of alcohol. Aliment Pharmacol Ther 2007; 26: 283-90. (Among 156 patients randomized to acetaminophen [4 g/day] or placebo for 10 days with liver tests at 0, 4 and 11 days, ALT elevations occurred in ~20% of acetaminophen treated patients; mostly <3 times ULN, only 1 >3 times ULN. On rechallenge, all redeveloped ALT elevations; no follow up). 17593074
Kc S. Acute liver failure caused by hepatitis E virus and paracetamol. JNMA J Nepal Med Assoc 2007; 46: 74-6. (45 year old man developed fatigue and body aches and took 4 g of acetaminophen for 2 days developing jaundice, stupor and coma [bilirubin 11.3 mg/dL, ALT 580 U/L, Alk P 406 U/L, IgM anti-HEV positive]; given N-acetylcysteine and recovered; authors raise issue of whether acetaminophen worsened course of acute hepatitis E). 18094741
Olosová, Lásová, Zaoral T, Bakhtary A. [The use of paracetamol in children--not just a drug but also a poison] Cas Lek Cesk 2007; 146: 401-5; discussion 405-6. Czech. 1749125
Satirapoj B, Lohachit P, Ruamvang T. Therapeutic dose of acetaminophen with fatal hepatic necrosis and acute renal failure. J Med Assoc Thai 2007; 90: 1244-7. (33 year old woman developed fatal acute liver failure while on therapeutic doses of acetaminophen [bilirubin 12.5 mg/dL, ALT 4640 U/L, creatinine 5.2 mg/dL]). 17624227
Schmidt LE, Larsen FS. MELD score as a predictor of liver failure and death in patients with acetaminophen-induced liver injury. Hepatology 2007; 45: 789-96. (MELD scores were reasonably predictive of hepatotoxicity and acute liver failure from acetaminophen, but not of survival). 17326205
Thomas MB, Moran N, Smart K, Crean S. Paracetamol overdose as a result of dental pain requiring medical treatment - two case reports. Br Dent J 2007; 203: 25-8. (Woman and man, both 20 years old, developed signs of overdose after taking excessive doses of acetaminophen [250-428 mg/kg] because of severe tooth pain; liver injury was mild and rapidly reversed). 17632482
Tokatli A, Kalkanoglu-Sivri HS, Yüce A, Coskun T. Acetaminophen-induced hepatotoxicity in a glutathione synthetase-deficient patient. Turk J Pediatr 2007; 49: 75-6. (Abstract: Nine month old girl with oxoprolinuria presented with metabolic acidosis but normal ALT levels after acetaminophen; probably unrelated). 17479648
Larson AM. Acetaminophen hepatotoxicity. Clin Liver Dis 2007; 11: 525-48. (Review of mechanisms and management of acetaminophen hepatotoxicity). 17723918
Wei G, Bergquist A, Broomé, Lindgren S, Wallerstedt S, Almer S, Sangfelt P, et al. Acute liver failure in Sweden: etiology and outcome. J Intern Med 2007; 262: 393-401. (Retrospective study of 279 patients presenting with acute liver failure during 10 years at 10 medical centers in Sweden; 118 [48%] were due to acetaminophen with spontaneous survival in 83%, transplantation in 5%, and death in 12%). 17697161
Kuffner EK, Green JL, Bogdan GM, Knox PC, Palmer RB, Heard K, Slattery JT, et al. The effect of acetaminophen (four grams a day for three consecutive days) on hepatic tests in alcoholic patients - a multicenter randomized study. BMC Medicine 2007; 5: 1-9. (443 subjects entering alcohol rehab program were randomized to acetaminophen [4 g/day] or placebo for 3 days; ALT levels rose slightly but similarly in acetaminophen and placebo recipients). 17537264
Hawkins LC, Edwards JN, Dargan PI. Impact of restricting paracetamol pack sizes on paracetamol poisoning in the United Kingdom: a review of the literature. Drug Saf 2007; 30: 465-79. (1998 legislation in UK restricted acetaminophen packaging and sales; 17 publications reviewed studies of effects of this legislation, many of which had conflicting results). 17536874
Amar PJ, Schiff ER. Acetaminophen safety and hepatotoxicity--where do we go from here? Expert Opin Drug Saf 2007; 6: 341-55. (Review with annotated references on acetaminophen hepatotoxicity). 17688378
Spiller HA, Sawyer TS. Impact of activated charcoal after acute acetaminophen overdoses treated with N-acetylcysteine. J Emerg Med 2007; 33: 141-4. (Retrospective analysis of reports of acetaminophen overdose; deaths were less common in those receiving both N-acetylcysteine [NAC] and activated charcoal [0.5%] compared to NAC alone [0.8%], but comparisons were not controlled for timing or severity). 17692765
Walls L, Baker CF, Sarkar S. Acetaminophen-induced hepatic failure with encephalopathy in a newborn. J Perinatol 2007; 27: 133-5. (4 day old infant admitted with renal and hepatic failure [bilirubin 9 mg/dl, ALT 978 U/L, protime 52 sec] after being given acetaminophen by parents for 3 days for circumcision pain; recovered with support and N-acetylcysteine infusions). 17262050
Ali FM, Boyer EW, Bird SB. Estimated risk of hepatotoxicity after an acute acetaminophen overdose in alcoholics. Alcohol 2008; 42: 213-8. (Calculated risk of hepatotoxicity after acetaminophen overdose using regression model arguing for a lower threshold for toxicity in abstinent alcoholics). 18358677
Allegaert K, Rayyan M, De Rijdt T, Van Beek F, Naulaers G. Hepatic tolerance of repeated intravenous paracetamol administration in neonates. Paediatr Anaesth 2008; 18: 388-92. (Intravenous acetaminophen is used in neonates for treatment of pain; in a retrospective analysis of liver tests before, during and after 1-4 days; among 2360 administrations in 189 children, no significant increases in ALT or AST found). 18384338
Carey EJ, Vargas HE, Douglas DD, Balan V, Byrne TJ, Harrison ME, Rakela J. Inpatient admissions for drug-induced liver injury: results from a single center. Dig Dis Sci 2008; 53: 1977-82. (Analysis of 40 cases of drug induced liver disease admitted to a single referral center over 8 year period; 27 were acetaminophen related, 1/3rd of which were unintentional [bilirubin 1.9-11.7 mg/dL, ALT 230-4422 U/L, Alk P 99-203 U/L], 6 fatal). 18392678
Grieco A, Miele L, Forgione A, Ragazzoni E, Vecchio FM, Gasbarrini G. Mild hepatitis at recommended doses of acetaminophen in patients with evidence of constitutionally enhanced cytochrome P450 system activity. J Clin Pharm Ther 2008; 33: 315-20. (37 year old woman and 57 year old man on 2 and 4 g of acetaminophen daily had ALT elevations [200 and 281 U/L] without symptoms or jaundice, resolving with stopping therapy; liver biopsies showed mild portal inflammation and minimal focal necrosis; antipyrine clearance testing suggested these patients had increased metabolism of acetaminophen through P450 system). 18452419
Hamwi I, Picksak G, Stichtenoth DO. [Accidental acetaminophen overdose] Med Monatsschr Pharm 2008; 31: 224-5. German. (Abstract: stresses importance of high doses of acetaminophen in causing unintentional hepatotoxicity). 18661913
Pearce B, Grant IS. Acute liver failure following therapeutic paracetamol administration in patients with muscular dystrophies. Anaesthesia 2008; 63: 89-91. (Two men, ages 20 and 42 years, with muscular dystrophy in ICU for respiratory failure were given acetaminophen [4 g daily] and developed acute liver failure within 3 days [bilirubin 19.4 and 7.3 mg/dL, ALT 2267 and 3850 U/L, prolonged INR]; both recovered; authors hypothesize that muscular dystrophy may be a risk factor). 18086077
Saviuc P, Danel V. [Acute acetaminophen overdose] Rev Prat 2008; 58: 861-5. French. (Review article on management of acetaminophen overdose). 18630824
Waring WS, Robinson OD, Stephen AF, Dow MA, Pettie JM. Does the patient history predict hepatotoxicity after acute paracetamol overdose? QJM 2008; 101: 121-5. (Prospective study of 987 patients with acetaminophen overdose, found patient history of amount taken was a partially reliable marker of subsequent liver injury; if ingestion was >12 g, 32% had hepatotoxicity; if <12 g, 3.2%). 18180256
Waring WS, Robinson OD, Stephen AF, Dow MA, Pettie JM. Serum urea concentration and the risk of hepatotoxicity after paracetamol overdose? QJM 2008; 101: 359-363. (Analysis of 1191 patients with acetaminophen overdose; baseline urea values did not predict development of hepatotoxicity, although urea values tended to be low in those admitting to chronic alcohol use). 18334496
James LP, Capparelli EV, Simpson PM, Letzig L, Roberts D, Hinson JA, Kearns GL, et al.; Network of Pediatric Pharmacology Research Units, National Institutes of Child Health and Human Development. Acetaminophen-associated hepatic injury: evaluation of acetaminophen protein adducts in children and adolescents with acetaminophen overdose. Clin Pharmacol Ther 2008; 84: 684-90. (Acetaminophen adducts were measured in 157 children presenting with overdose; peak adduct levels correlated with AST and ALT levels, time after overdose, and nomogram risk). 18923390
Bartels S, Sivilotti M, Crosby D, Richard J. Are recommended doses of acetaminophen hepatotoxic for recently abstinent alcoholics? A randomized trial. Clin Toxicol 2008; 46: 243-9. (Randomized controlled trial of acetaminophen [4 g/day for 4 days] vs placebo in 52 patients in an alcohol withdrawal program, found no differences in ALT or AST levels over 5 days). 18344107
Polson J, Wians FH Jr, Orsulak P, Fuller D, Murray NG, Koff JM, Khan AI, et al.; Acute Liver Failure Study Group. False positive acetaminophen concentrations in patients with liver injury. Clin Chim Acta 2008; 391: 24-30. (Assessment of 6 different assays for plasma acetaminophen levels found frequent, but low level false positive results using colorimetric, but not immunoassays; probably due to bilirubin). 18279672
Murray KF, Hadzic N, Wirth S, Bassett M, Kelly D. Drug-related hepatotoxicity and acute liver failure. J Pediatr Gastroenterol Nutr 2008; 47: 395-405. (Review of drug induced acute liver failure in children; among 348 cases in Pediatric ALF Study, 14% were due to acetaminophen [94% spontaneous survival without transplant] and 5% to other medications [only 36% spontaneous survival]). 18852631
Smith SW, Howland MA, Hoffman RS, Nelson LS. Acetaminophen overdose with altered acetaminophen pharmacokinetics and hepatotoxicity associated with premature cessation of intravenous N-acetylcysteine therapy. Ann Pharmacother 2008; 42: 1333-9. (78 year old man took 48 g of acetaminophen and was started on iv N-acetylcysteine [NAC] within 5 hours; serum acetaminophen levels fell, but then rose 12-24 hours after the 21-hour NAC infusion was stopped with subsequent marked rise in ALT [5621 U/L]; NAC continued for 10 more days and patient survived). 18628444
Myers RP, Shaheen AA, Li B, Dean S, Quan H. Impact of liver disease, alcohol abuse, and unintentional ingestions on the outcomes of acetaminophen overdose. Clin Gastroenterol Hepatol 2008; 6: 918-25 (Among 1543 patients with acetaminophen overdose seen between 1995-2004 followed in a Canadian health care region, 4.5% developed hepatotoxicity; in multivariate analysis risk factors for liver injury were underlying liver disease, unintentional overdose and alcohol abuse). 18486561
Doyon S, Klein-Schwartz W. Hepatotoxicity despite early administration of intravenous N-acetylcysteine for acute acetaminophen overdose. Acad Emerg Med 2009; 16: 34-9. (Retrospective analysis of 77 patients with acetaminophen overdose receiving 21 hours of iv N-acetylcysteine starting 1-8 hours after ingestion, 7 patients [9%] had acetaminophen detectable in serum or elevated ALT levels at end of therapy, one of whom died and one underwent liver transplant for acute liver failure, suggesting that therapy should be prolonged for some patients). 19007345
Majlesi N, Olsen A, Krishnan GP, Olsen D, Nelson L. Hepatotoxicity despite early administration of intravenous N-acetylcysteine for acute acetaminophen overdose. Acad Emerg Med 2009; 16: 574; author reply 575. (Letter in response to Doyon [2009] raising issue of unusual finding of late rise in levels of acetaminophen and the possibility of re-ingestion). 19426297
Cooper SC, Aldridge RC, Shah T, Webb K, Nightingale P, Paris S, Gunson BK, et al. Outcomes of liver transplantation for paracetamol(acetaminophen)-induced hepatic failure. Liver Transpl 2009; 15: 1351-7. (Among 858 patients with acute liver injury from acetaminophen seen in a UK center between 1989 and 207, 60 [7%] underwent liver transplantation of whom 73% survived to discharge and 58% survived long term, these rates being lower than for transplantation for chronic liver disease or other forms of acute liver failure). 19790165
Suzuki A, Yuen N, Walsh J, Papay J, Hunt CM, Diehl AM. Co-medications that modulate liver injury and repair influence clinical outcome of acetaminophen-associated liver injury. Clin Gastroenterol Hepatol 2009; 7: 882-8. (Analysis of acetaminophen-induced liver injury from the FDA Adverse Event Reporting System comparing fatal [n=2512] to non-fatal [n=3874] cases found higher rates of alcohol use, but lower rates of statin and nonsteroid antiinflammatory drug use among fatal cases). 19362607
Myers RP, Shaheen AA. Hepatitis C, alcohol abuse, and unintentional overdoses are risk factors for acetaminophen-related hepatotoxicity. Hepatology 2009; 49: 1399-400. (Analysis of database of 42,718 hospitalizations for acetaminophen overdose, of which 1.7% had hepatitis C who had a higher rate of hepatotoxicity [16.7% vs 4.5%] than noninfected overdose patients). 19330871
Kubic A, Burda AM, Bockewitz E, Wahl M. Hepatotoxicity in an infant following supratherapeutic dosing of acetaminophen for twenty-four hours. Semin Diagn Pathol 2009; 26: 7-9. (7 month old boy was given higher than recommended dose of acetaminophen [234 mg/kg/24 hours: 1.8 g] and presented with vomiting [bilirubin 0.3 mg/dL, ALT 907 U/L, AST 1339 U/L, Alk P 205 U/L], responding to iv N-acetylcysteine for 37 hours with rapid improvement and had normal enzyme levels 10 days later). 19292023
Betten DP, Burner EE, Thomas SC, Tomaszewski C, Clark RF. A retrospective evaluation of shortened-duration oral N-acetylcysteine for the treatment of acetaminophen poisoning. J Med Toxicol 2009; 5: 183-90. (Retrospective analysis of outcome of shortened courses of oral N-acetylcysteine for acetaminophen overdose based upon analysis of 1932 cases reported to the California Poison Control System between 1999-2003, follow up finding no evidence of deaths from liver failure in those with early discontinuation). 19876849
Miller AL. Liver damage from chronic acetaminophen dosing is dangerous, but not the only risk. Altern Med Rev 2009; 14: 322-3. (Editorial discussing role of acetaminophen in causing ALT elevations, but also affecting immune system and possibly causing autism). 20030459
Jickling G, Heino A, Ahmed SN. Acetaminophen toxicity with concomitant use of carbamazepine. Epileptic Disord 2009; 11: 329-32. (34 year old man on long term carbamazepine developed abdominal pain 2 weeks after starting 2.0-2.5 g of acetaminophen daily [bilirubin not given, ALT 9101 U/L], enzymes falling to normal within 2 weeks with N-acetylcysteine and prednisone therapy). 19995690
Yarema MC, Johnson DW, Berlin RJ, Sivilotti ML, Nettel-Aguirre A, Brant RF, Spyker DA, et al. Comparison of the 20-hour intravenous and 72-hour oral acetylcysteine protocols for the treatment of acute acetaminophen poisoning. Ann Emerg Med 2009; 54: 606-14. (Retrospective comparison of 20 hour intravenous vs 72 hour oral regimen of N-acetylcysteine [NAC] for acetaminophen overdose in 4048 patients, found rates of hepatotoxicity [AST or ALT >1000 U/L] of 13.9% vs 15.8%. 1 patient underwent transplant with iv regimen [20 hours] and 3 patients died with oral regimen [19-24 hours]; iv regimen may have been superior for early and oral for late cases; anaphylactic reaction to iv NAC in 7.1%). 19556028
Gupta AK, Su MK, Greller HA, Lee DC, Chan GM. IV versus oral N-acetylcysteine. Ann Emerg Med 2009; 54: 857-8; author reply 858-9. (Letter in response to Yarema [2009] questioning whether AST elevations should be used as an endpoint in assessing efficacy of N-acetylcysteine regimens). 19942075
Bond GR. Is the oral acetylcysteine protocol the best treatment for late-presenting acetaminophen poisoning? Ann Emerg Med 2009; 54: 615-7. (Editorial regarding Yarema [2009] discussing the shortcomings of data on the optimal regimen of N-acetylcysteine therapy for acetaminophen overdose). 19695740
Traynor K. FDA's acetaminophen meeting sparks confusion, uncertainty. Am J Health Syst Pharm 2009; 66: 1422, 1425-6. (News article on 2009 FDA meeting on the safety of acetaminophen and possible steps to decrease the amount in prescription and nonprescription products). 19666995
Kuehn BM. FDA focuses on drugs and liver damage: labeling and other changes for acetaminophen. JAMA 2009; 302: 369-71. (News article on FDA initiative to reduce acetaminophen associated liver injury, reports of which increased from 89 in 1995 to 404 in 2005). 19622807
Acetaminophen safety - deja vu. Med Lett Drugs Ther 2009; 51 (1316): 53-4, 56. (Reprint of a brief overview of acetaminophen effectiveness and safety from 2002). 19590488
Levi N, Bastuji-Garin S, Mockenhaupt M, Roujeau JC, Flahault A, Kelly JP, Martin E, et al. Medications as risk factors of Stevens-Johnson syndrome and toxic epidermal necrolysis in children: a pooled analysis. Pediatrics 2009; 123: e297-304. (Among 80 cases of SJS/TEN in children [<15 years] identified in 2 large prospective databases from Europe, the most commonly implicated drugs were antibiotics, antiepileptics and NSAIDs, but 24 children [37%] were exposed to acetaminophen in the week before onset compared to 7% [11/216] controls). 19153164
Trujillo C, Gago C, Ramos S. Stevens-Jonhson syndrome after acetaminophen ingestion, confirmed by challenge test in an eleven-year-old patient. Allergol Immunopathol (Madr) 2010; 38: 99-100. (11 year old boy developed rash with target-like bullae followed by SJS 3 days after starting acetaminophen for a cold, having previously tolerated it; after recovery he redeveloped skin rash within 48 hours of re-exposure [no liver test results provided]). 19875224
Duh MS, Vekeman F, Korves C, Lefebvre P, Dial E, Latremouille-Viau D, Wei RS, et al. Risk of hepatotoxicity-related hospitalizations among patients treated with opioid/acetaminophen combination prescription pain medications. Pain Med 2010; 11: 1718-25. (Retrospective cohort study examining insurance claims; found no increased risk of hospitalization due to opioid/acetaminophen combination). 21044262
Green TJ, Sivilotti ML, Langmann C, Yarema M, Juurlink D, Burns MJ, Johnson DW. When do the aminotransferases rise after acute acetaminophen overdose? Clin Toxicol (Phila) 2010; 48: 787-92. (Analysis of early changes in ALT levels in 94 cases of acetaminophen overdose with liver injury from a Canadian registry showed that ALT levels were usually elevated within 24 hours of ingestion and rose above 1,000 U/L by 24 to 48 hours). 20969501
Jepsen P, Schmidt LE, Larsen FS, Vilstrup H. Long-term prognosis for transplant-free survivors of paracetamol-induced acute liver failure. Aliment Pharmacol Ther 2010; 32: 894-900. (Among 641 patients who survived after acetaminophen overdose with liver injury in Denmark, rates of long term survival were similar in those who had acute liver failure compared to those with milder injury; none died of cirrhosis or liver failure, suicide was frequent). 20735774
Lee WM. The case for limiting acetaminophen-related deaths: smaller doses and unbundling the opioid-acetaminophen compounds. Clin Pharmacol Ther 2010; 88: 289-92. (Since 2000, acetaminophen has accounted for 38-53% of cases of acute liver failure in the United States and half of cases were unintentional overdose; discussion of regulatory approaches to decreasing this problem). 20725075
Heard KJ, Green JL, Dart RC. Serum alanine aminotransferase elevation during 10 days of acetaminophen use in nondrinkers. Pharmacotherapy 2010; 30: 818-22. (Among 24 healthy volunteers given acetaminophen [4 g daily] for 10 days, 58% developed at least one ALT elevation, but all were mild [peak ~140 U/L], transient, and not associated with symptoms or bilirubin elevations). 20653358
Devarbhavi H, Dierkhising R, Kremers WK, Sandeep MS, Karanth D, Adarsh CK. Single-center experience with drug-induced liver injury from India: causes, outcome, prognosis, and predictors of mortality. Am J Gastroenterol 2010; 105: 2396-404. (Among 313 cases of drug induced liver injury seen over a 12 year period at a large hospital in Bangalore, India, <1% were attributed to acetaminophen). 20648003
Bernal W, Auzinger G, Dhawan A, Wendon J. Acute liver failure. Lancet 2010; 376(9736): 190-201. (Review describes acute liver failure caused by acetaminophen as "hyperacute", with rapid onset of encephalopathy, severe coagulopathy, mild to moderate jaundice and high rate of survival without transplantation; accounting for 36-57% of cases in UK, US, Australia and Sweden, but only 2% in Spain and <1% in India, Pakistan and the Sudan). 20638564
Albertson TE, Walker VM Jr, Stebbins MR, Ashton EW, Owen KP, Sutter ME. A population study of the frequency of high-dose acetaminophen prescribing and dispensing. Ann Pharmacother 2010; 44: 1191-5. (Analysis of Medicaid pharmacy claims over a 1 year period in California found 5.9% of beneficiaries were potentially exposed to >4 g and some >16 g of acetaminophen daily). 20551297
Livshits Z, Hoffman RS. Comment: a population study of the frequency of high-dose acetaminophen prescribing and dispensing. Ann Pharmacother 2010; 44: 1856. (Letter in response to Albertson [2010] raising issue of whether liver injury arises as a result of standard [up to 4 g/day] or only with higher doses). 20959504
Dart RC, Green JL, Kuffner EK, Heard K, Sproule B, Brands B. The effects of paracetamol (acetaminophen) on hepatic tests in patients who chronically abuse alcohol - a randomized study. Aliment Pharmacol Ther 2010; 32: 478-86. (Among 142 newly abstinent, alcoholic subjects given acetaminophen [4 g daily] or placebo for 5 days, mean ALT levels rose minimally in both acetaminophen [48 to 62 U/L] and placebo [47 to 49 U/L] groups, while bilirubin levels fell and INR values were stable). 20491750
Michna E, Duh MS, Korves C, Dahl JL. Removal of opioid/acetaminophen combination prescription pain medications: assessing the evidence for hepatotoxicity and consequences of removal of these medications. Pain Med 2010; 11: 369-78. (Review of the literature on the role of opioid/acetaminophen combinations in causing hepatotoxicity concluded "there is no reliable information from which we can draw conclusions about the absolute or relative risk of these medications", which led authors to argue against regulatory restriction of this combination). 20447306
Hendrickson RG, McKeown NJ, West PL, Burke CR. Bactrian ("double hump") acetaminophen pharmacokinetics: a case series and review of the literature. J Med Toxicol 2010; 6: 337-44. (Three patients, 2 women and one boy, ages 38, 25 and 16 years, were seen soon after large acetaminophen overdoses [65, 26 and 100 g] and found to have a second rise in serum acetaminophen levels at 37-42 hours with subsequent liver injury [peak ALT 2351, 2236 and 10,832 U/L at 97, 109 and 91 hours], all received N-acetylcysteine and all survived). 20446076
Karvellas CJ, Safinia N, Auzinger G, Heaton N, Muiesan P, O'Grady J, Wendon J, et al. Medical and psychiatric outcomes for patients transplanted for acetaminophen-induced acute liver failure: a case-control study. Liver Int 2010; 30: 826-33. (Outcome after liver transplantation was similar for patients with acetaminophen- vs non-acetaminophen induced acute liver failure, but 2 of 36 acetaminophen cases subsequently reattempted suicide, one successfully). 20408947
Barritt AS 4th, Lee J, Hayashi PH. Detective work in drug-induced liver injury: sometimes it is all about interviewing the right witness. Clin Gastroenterol Hepatol 2010; 8: 635-7. (4 patients with drug induced liver injury were misdiagnosed because the drug was not mentioned or acknowledged in the initial medical history; alfuzosin, acetaminophen and, in two, amoxicillin/clavulanate). 20363371
Zyoud SH, Awang R, Sulaiman SA, Al-Jabi SW. Association between gastrointestinal manifestations following acetaminophen poisoning and outcome in 291 acetaminophen poisoning patients. Pharmacoepidemiol Drug Saf 2010; 19: 511-7. (Among 291 patients with acetaminophen overdose seen over a 5 year period, 77% developed gastroinestinal manifestations [nausea, pain, diarrhea] which were associated with higher doses, longer latency and more renal and hepatic complications, but no patient died). 20333776
Gregory B, Larson AM, Reisch J, Lee WM; Acute Liver Failure Study Group. Acetaminophen dose does not predict outcome in acetaminophen-induced acute liver failure. J Investig Med 2010; 58: 707-10. (Analysis of estimated dose of acetaminophen with risk of acute liver failure after intentional overdose found that the dose estimates did not correlate well with severity or outcome). 20305573
Graham GG, Day RO, Graudins A, Mohamudally A. FDA proposals to limit the hepatotoxicity of paracetamol (acetaminophen): are they reasonable? Inflammopharmacology 2010; 18: 47-55. (Discussion of the options proposed by the FDA for limiting the hepatotoxicity of acetaminophen). 20213329
Bateman DN, Dear J. Medicine, poison, and mystic potion: a personal perspective on paracetamol Louis Roche lecture, Stockholm, 2009. Clin Toxicol (Phila) 2010; 48: 97-103. (Review of the history of diagnosis and management of acetaminophen overdose). 20199128
Winnike JH, Li Z, Wright FA, Macdonald JM, O'Connell TM, Watkins PB. Use of pharmaco-metabonomics for early prediction of acetaminophen-induced hepatotoxicity in humans. Clin Pharmacol Ther 2010; 88: 45-51. (Analysis of urinary metabonomic profiles in healthy volunteers given acetaminophen [4 g daily] for 7 days [Watkins 2006] identified N-acetyl paraquinone imine [NAPQ] metabolites that predicted who would develop liver injury before the actual onset). 20182423
Lavonas EJ, Reynolds KM, Dart RC. Therapeutic acetaminophen is not associated with liver injury in children: a systematic review. Pediatrics 2010; 126: e1430-44. (Systematic review of literature on acetaminophen hepatotoxicity in children receiving therapeutic doses [<75 mg/kg/day]; no instance of clinically apparent liver injury was reported in defined population studies; but 22 published case reports were identified, although on re-review only 9 were considered probable). 21098156
Shivbalan S, Sathiyasekeran M, Thomas K. Therapeutic misadventure with paracetamol in children. Indian J Pharmacol 2010; 42: 412-5. (Six infants, ages 6 weeks to 3 years, were given excessive doses of acetaminophen [100-367 mg/k/day] and were treated with N-acetylcysteine, 3 had ALT elevations [1026, 529 and 569 U/L], 5 recovered and 1 [who also had dengue fever] died of multiorgan failure). 21189918
Claridge LC, Eksteen B, Smith A, Shah T, Holt AP. Acute liver failure afteradministration of paracetamol at the maximum recommended daily dose in adults. BMJ 2010; 341: c6764. (43 year old man with Crohn disease given acetaminophen [4 g daily] for 4 days developed acute liver failure [AST 12,769 U/L, INR 9.1] and died 12 days later despite prompt therapy with N-acetylcysteine [NAC]; 32 year old woman with alcoholism given acetaminophen [4 g daily] for 3 days developed acute liver failure [AST 7116 U/L, INR 3.2] and recovered after NAC therapy). 21127120
Claridge LC, Eksteen B, Smith A, Shah T, Holt AP. [Acute liver failure after administration of paracetamol at the maximum recommended daily dose in adults]. Praxis (Bern 1994) 2011; 100: 923-6. German. (German language version of Claridge [2010]). 21792808
Haga C, Muan B, Cheung M, Lyngra M, Strømsæther CE, Lutro O, Andrew E. [Paracetamol poisonings after the lifting of the place of sale restriction]. Tidsskr Nor Laegeforen 2011; 131: 2115-8. Norwegian. (Analysis of a national poison registry in Norway between 2001 and 2006 found no increase in hospitalizations for acetaminophen poisonings despite national restrictions on its purchase being lifted in 2003). 22048206
Starkey Lewis PJ, Dear J, Platt V, Simpson KJ, Craig DG, Antoine DJ, French NS, et al. Circulating microRNAs as potential markers of human drug-induced liver injury. Hepatology 2011; 54: 1767-76. (Liver associated micro-RNA levels [miR-122 and miR-192] were elevated in cases of acute liver injury due to acetaminophen and other causes compared to controls; miR-122 levels correlated best with ALT elevations). 22045675
Mort JR, Shiyanbola OO, Ndehi LN, Xu Y, Stacy JN. Opioid-paracetamol prescription patterns and liver dysfunction: a retrospective cohort study in a population served by a US health benefits organization. Drug Saf 2011; 34: 1079-88. (Analysis of data from 4.8 million health beneficiaries found 5.3 million prescriptions for opioid-acetaminophen combinations, 19% of which exceeded the recommended maximal daily acetaminophen dose of 4 g). 21981435
Palmer KA, Shane R. Care needed with i.v. acetaminophen. Am J Health Syst Pharm 2011; 68: 1775-6. (Letter on the potential of making errors in dosing of intravenous acetaminophen and the need for care). 21930633
Chomchai S, Chomchai C, Anusornsuwan T. Acetaminophen psi parameter: a useful tool to quantify hepatotoxicity risk in acute acetaminophen overdose. Clin Toxicol (Phila) 2011; 49: 664-7. (Analysis of whether the psi parameter [acetminophen level 4 hours after ingestion and time to start of N-acetylcysteine] was predictive of hepatotoxicity). 21819286
Li C, Martin BC. Trends in emergency department visits attributable to acetaminophen overdoses in the United States: 1993-2007. Pharmacoepidemiol Drug Saf 2011; 20: 810-8. (Estimated rates of emergency department visits due to acetaminophen overdose decreased from 21 to 15 per 100,000 person-years between 1993 and 2007 and accounted for 44-56,000 visits yearly). 21796717
Sabaté M, Ibáñez L, Pérez E, Vidal X, Buti M, Xiol X, Mas A, et al. Paracetamol in therapeutic dosages and acute liver injury: causality assessment in a prospective case series. BMC Gastroenterol 2011; 11: 80. (In a population-based study conducted in Spain between 1993 and 2000, 32 of 126 cases of acute liver injury were identified in patients taking "therapeutic" doses of acetaminophen, but only 4 cases were considered probably and 3 possibly due to acetaminophen using the RUCAM scoring system, yielding an population based incidence of 10 per million acetaminophen users). 21762481
Clement C, Scala-Bertola J, Javot L, Royer-Morrot MJ, Gillet P, Trechot P, Petitpain N, et al. Misuse of acetaminophen in the management of dental pain. Pharmacoepidemiol Drug Saf 2011; 20: 996-1000. (During a 9 month period, 13 cases of unintentional acetaminophen overdose [71-842 mg/kg/24 hr] in dental patients were reported to a French Pharmacovigilance Center; 7 subjects had symptoms, 4 had ALT elevations, 4 received NAC, but none had acute liver failure or died). 21726014
Brusilow SW, Cooper AJ. Encephalopathy in acute liver failure resulting from acetaminophen intoxication: new observations with potential therapy. Crit Care Med 2011; 39: 2550-3. (22 year old woman with an acetaminophen overdose [15 g] presented 36 hours later with nausea [biliurbin 12.9 mg/dL, ALT 6710 U/L, ammonia >200 microM], but went into coma at 72 hours as ammonia and ALT levels fell suggesting that brain glutamine rather than ammonia was responsible for coma). 21705899
King JP, Davis TC, Bailey SC, Jacobson KL, Hedlund LA, Di Francesco L, Parker RM, et al. Developing consumer-centered, nonprescription drug labeling a study in acetaminophen. Am J Prev Med 2011; 40: 593-8. (Interviews of 6 consumer focus groups found only 31% of participants knew that Tylenol contained acetaminophen and many had a poor understanding of "active ingredient"; authors recommended use of icons for portraying the active ingredient and maximum dose). 21565649
Mitchell SJ, Hilmer SN, Murnion BP, Matthews S. Hepatotoxicity of therapeutic short-course paracetamol in hospital inpatients: impact of ageing and frailty. J Clin Pharm Ther 2011; 36: 327-35. (Among 71 hospitalized patients treated with acetaminophen [3-4 g/day for at least 5 days], mean ALT levels at 5 days were higher in younger patients and in older patients who were not frail, but specific results not given). 21545612
Ferner RE, Dear JW, Bateman DN. Management of paracetamol poisoning. BMJ 2011; 342: 2218. (Review of management of acetaminophen overdose). 21508044
Heard KJ, Green JL, James LP, Judge BS, Zolot L, Rhyee S, Dart RC. Acetaminophen-cysteine adducts during therapeutic dosing and following overdose. BMC Gastroenterol 2011; 11: 20. (Most subjects participating in clinical trials of therapeutic doses of acetaminophen had detectable levels of cysteine adducts in serum, but always <1.1 nmol/mL, while subjects with severe hepatotoxicity [ALT >1000 U/L] usually had levels >1.1 nmol/mL). 21401949
Alhelail MA, Hoppe JA, Rhyee SH, Heard KJ. Clinical course of repeated supratherapeutic ingestion of acetaminophen. Clin Toxicol (Phila) 2011; 49: 108-12. (Among 503 acetaminophen overdose cases treated with N-acetylcysteine, 119 [24%] were considered due to repeated supratherapeutic ingestion of whom 41 [34%] developed ALT >1000 U/L, 4 died and 2 had a liver transplant; hepatotoxicity occurred only in those with raised ALT at presentation [lowest 252 U/L] and was more frequent in those with a history of alcoholicsm, viral hepatitis, and INR above 1.5 or creatinine 1.3 mg/dL at presentation). 21370947
Heard K. Asymptomatic alanine aminotransferase elevations with therapeutic doses of acetaminophen. Clin Toxicol (Phila) 2011; 49: 90-3. (Editorial on frequency and possible significance of ALT elevations occurring during acetaminophen therapy as identified in several prospective studies; virtually all cases were self limiting, asymptomatic and without accompanying bilirubin elevations). 21370944
Offerman SR. The clinical management of acetaminophen poisoning in a community hospital system: factors associated with hospital length of stay. J Med Toxicol 2011; 7: 4-11. (Retrospective analysis of 435 cases of acetaminophen overdose managed in the Northern California Kaiser Permanente system between 2003 and 2008 found similar hospital length of stay with iv as with oral N-acetylcysteine therapy; 4 patients died, none underwent liver transplantation). 20857257
Khandelwal N, James LP, Sanders C, Larson AM, Lee WM; and the Acute Liver Failure Study Group. Unrecognized acetaminophen toxicity as a cause of indeterminate acute liver failure. Hepatology 2011; 53: 567-76. ( Among 110 patients with acute liver failure of unknown cause, 20 [18%] had acetaminophen-cysteine adducts above 1.0 nmol/mL, all of whom had other features suggestive of acetaminophen injury [young age, female sex, ALT > 1000 U/L, modest bilirubin elevations, high rate of spontaneous survival]). 21274877
Claridge LC. Detection of acetaminophen-cysteine adducts in cases of indeterminate liver failure is not diagnostic of intentional overdose. Hepatology 2011; 54: 746-7. (Letter in response to Khandelwal [2011] suggesting that all cases of indeterminate acute liver failure should be treated with N-acetylcysteine). 21360569
Bisschops LA, Bisschops WA, Vroegop MP, van Rossum LK, Kramers C. [Intentional paracetamol intoxication in children]. Ned Tijdschr Geneeskd 2011; 155: A2132. Dutch. (Review of management of acetaminophen overdose in children). 21262016
Ceelie I, James LP, Gijsen V, Mathot RA, Ito S, Tesselaar CD, Tibboel D, Koren G, de Wildt SN. Acute liver failure after recommended doses of acetaminophen in patients with myopathies. Crit Care Med 2011; 39: 678-82. (Two girls, ages 12 and 17, with myopathies were treated with recommended doses of rectal acetaminophen and developed acute liver failure [AST >2000 U/L, acetaminophen-cysteine adducts >1 nmol/mL], given N-acetylcysteine, one died and one survived; suggested an increased susceptibility of patients with myopathy). 21242792
Craig DG, Bates CM, Davidson JS, Martin KG, Hayes PC, Simpson KJ. Overdose pattern and outcome in paracetamol-induced acute severe hepatotoxicity. Br J Clin Pharmacol 2011; 71: 273-82. (Among 938 patients with severe liver injury admitted to a Scottish Transplant center over an 18 year period, 663 were attributed to acetaminophen of which 75% were intentional, 17% unintentional, 8% unknown; the unintentional cases being older and having a lower spontaneous survival rate [57% vs 74%]). 21219409
Mehrpour O, Shadnia S, Sanaei-Zadeh H. Late extensive intravenous administration of N-acetylcysteine can reverse hepatic failure in acetaminophen overdose. Hum Exp Toxicol 2011; 30: 51-4. (18 year old man with acetaminophen overdose [34 g] presented with vomiting and jaundice 2 days later [ALT 870 U/L, bilirubin 10.3 mg/dL, INR 6], was given 6 days of iv N-acetylcysteine and survived). 20332167
Shah AD, Wood DM, Dargan PI. Understanding lactic acidosis in paracetamol (acetaminophen) poisoning. Br J Clin Pharmacol 2011; 71: 20-8. (Commentary on meaning of lactic acidosis in patients with acetaminophen overdose). 21143497
Beringer RM, Thompson JP, Parry S, Stoddart PA. Intravenous paracetamol overdose: two case reports and a change to national treatment guidelines. Arch Dis Child 2011; 96: 307-8. (Two infants, ages 5 and 6 months, were given a single incorrect dose of iv acetaminophen [75 and 90 rather than 15 mg/kg] and were given N-acetylcysteine, 1 developing liver injury [peak bilirubin 2.0 mg/dL, ALT 2819 U/L, INR 3.6], resolving within 6 days). 21127004
Klein-Schwartz W, Doyon S. Intravenous acetylcysteine for the treatment of acetaminophen overdose. Expert Opin Pharmacother 2011; 12: 119-30. (Review of the efficacy and safety of N-acetylcysteine for acetaminophen overdose suggests that standard regimen is adequate for uncomplicated cases with early presentation, but that extended courses may be better for high risk patients). 21126198
O'Connor ES, Schwarze ML, Kodner IJ, Keune JD. Surrogate decision making: a woman in fulminant liver failure after an acetaminophen overdose. Surgery 2011; 150: 1006-10. (Discussion of the ethical issues surrounding management of a woman with acute liver failure after acetaminophen overdose who is comatose and unable to provide consent for interventions including potentially life-saving liver transplantation). 22132422
Starkey Lewis PJ, Dear J, Platt V, Simpson KJ, Craig DG, Antoine DJ, French NS, et al. Circulating microRNAs as potential markers of human drug-induced liver injury. Hepatology 2011; 54: 1767-76. (Circulating miRNA-122 levels were elevated in patients with acute liver failure and particularly with acetaminophen overdose, with a higher dynamic range and more rapid recovery than ALT levels). 22045675
Zyoud SH, Awang R, Sulaiman SA. Reliability of the reported ingested dose of acetaminophen for predicting the risk of toxicity in acetaminophen overdose patients. Pharmacoepidemiol Drug Saf 2012; 21: 207-13. (Among 291 patients presenting within 24 hours of an acetaminophen overdose to a Malaysian hospital center, 97% of those reporting ingestion of >8 g had serum levels above the possible toxicity treatment line compared to only 3% of those reporting <8 g). 21812068
Dart RC, Rumack BH. Intravenous acetaminophen in the United States: iatrogenic dosing errors. Pediatrics 2012; 129: 349-53. (Review of the use and safety of iv acetaminophen [approved for use in the United States in 2011] and review of reports of 3 cases of dosing errors in children, only one of which was followed by liver injury and may not have been the cause). 22271694
Craig DG, Reid TW, Wright EC, Martin KG, Davidson JS, Hayes PC, Simpson KJ. The sequential organ failure assessment (SOFA) score is prognostically superior to the model for end-stage liver disease (MELD) and MELD variants following paracetamol (acetaminophen) overdose. Aliment Pharmacol Ther 2012; 35: 705-13. (Evaluation of two scoring systems [SOFA and MELD] for predicting acute liver failure and spontaneous survival in 138 patients with acetaminophen overdose). 22260637
Khawaja A, Shahab A, Hussain SA. Acetaminophen induced Steven Johnson syndrome-toxic epidermal necrolysis overlap. J Pak Med Assoc 2012; 62: 524-7. (40 year old woman took two doses of acetaminophen for fever and developed rash with oral and eye involvement evolving into severe SJS/TEN overlap [liver tests reported to be normal], ultimately recovery with corticosteroids, no rechallenge). 22755330
Zhou L, Maviglia SM, Mahoney LM, Chang F, Orav EJ, Plasek J, Boulware LJ, et al. Supratherapeutic dosing of acetaminophen among hospitalized patients. Arch Intern Med 2012; 172: 1721-8. (Analysis of electronic health records from 2 teriary care hospitals over a 6 month period found 14,411 patients who were exposed to acetaminophen, the dose exceeding 4 g daily in 955 [7%]). 23401887
Rodriguez Lopez M, Perez Saborido B, Pacheco Sanchez D, Asensio Diaz E, Labarga Rodriguez F, Martinez Diaz R, Gonzalo Martin M, et al. Transplantation for acute liver failure: report of results in the region of Castilla y Leon (Spain) after 10 years of activity. Transplant Proc 2012; 44: 2625-6. (among 325 patients undergoing liver transplantation at a single center in Spain between 2001-2011, 14 [4.3%] were done for acute liver failure, but none for acetaminophen overdose). 23146476
Ji P, Wang Y, Li Z, Doddapaneni S, Hertz S, Furness S, Sahajwalla CG. Regulatory review of acetaminophen clinical pharmacology in young pediatric patients. J Pharm Sci 2012; 101: 4383-9. (Review of the pharmacokinetics of acetaminophen in children as it relates to recommended doses: 10-15 mg/kg for children of 6 months to 12 years of age). 23073837
Marzilawati AR, Ngau YY, Mahadeva S. Low rates of hepatotoxicity among Asian patients with paracetamol overdose: a review of 1024 cases. BMC Pharmacol Toxicol 2012; 13: 8. (Among 1024 patients presenting with acetaminophen overdose during a 5 year period to 2 large public hospitals in Mayalsia, 124 [[12%] had mild and 73 [7%] severe hepatotoxicity [ALT >1000 U/L], but none died). 23021009
Bebarta VS, Shiner DC, Varney SM. A case of moderate liver enzyme elevation after acute acetaminophen overdose despite undetectable acetaminophen level and normal initial liver enzymes. Am J Ther 2014;21:382-4. (22 year old man had normal serum enzyme and no detectable acetaminophen in serum 16 hours after a suicidal overdose of 7.5-12.5 g, yet ALT levels subsequently rose peaking at ~405 U/L 2 days later, then falling rapidly). 23011168
Varney SM, Buchanan JA, Kokko J, Heard K. Acetylcysteine for Acetaminophen Overdose in Patients Who Weigh >100 Kg. Am J Ther 2012 Sep 24. [Epub ahead of print] (Analysis of a prospective study of iv vs oral acetylcysteine therapy of acetaminophen overdose identified 37 patients who weighed more than 100 kg of whom 34 received a weight-based dose, although recommendations are for a maximum dose based on a maximum weight of 100 kg [iv] or 110 kg [oral]). 23011167
Kaufman DW, Kelly JP, Rohay JM, Malone MK, Weinstein RB, Shiffman S. Prevalence and correlates of exceeding the labeled maximum dose of acetaminophen among adults in a U.S.-based internet survey. Pharmacoepidemiol Drug Saf 2012; 21: 1280-8. (An internet survey of 5649 persons regarding their understanding of the risks of acetaminophen found that 3618 used acetaminophen and 163 [4.5%] took more than 4 g daily at least once weekly, usually for chronic pain). 23001694
Goyal RK, Rajan SS, Essien EJ, Sansgiry SS. Effectiveness of FDA's new over-the-counter acetaminophen warning label in improving consumer risk perception of liver damage. J Clin Pharm Ther 2012; 37: 681-5. (Survey of 205 persons who were visiting a pharmacy regarding risks of acetaminophen found that new warning labels increased their assessment of risk). 22958105
Kane A, Mitchell SJ, Carroll PR, Matthews S, Hilmer SN. Characteristics of older and younger patients with suspected paracetamol toxicity. Australas J Ageing 2012; 31: 190-3. (Among 359 patients admitted to a large medical center in Sydney who had detectable serum acetaminophen levels, 50 were 20-30 years old [younger group] and 25 were 65 or above [older group], the older being more likely to have unintentional overdose [90% vs 29%] and abnormal ALT levels [42% vs 6%], but all recovered regardless of age). 22950592
Iorio ML, Cheerharan M, Kaufman SS, Reece-Stremtan S, Boyajian M. Acute liver failure following cleft palate repair: a case of therapeutic acetaminophen toxicity. Cleft Palate Craniofac J 2013; 50: 747-50. (8 month old boy underwent cleft palate repair and 3 days later was admitted with lethargy, seizures and acute hepatitis [bilirubin 3.1 mg/dL, ALT 12,885 U/L] which was attributed to acetaminophen [levels 83 mg/L] prescribed for post surgical pain). 22937760
Leung PS, Lam K, Kurth MJ, Coppel RL, Gershwin ME. Xenobiotics and autoimmunity: does acetaminophen cause primary biliary cirrhosis? Trends Mol Med 2012; 18: 577-82. (Hypothesis that high doses of acetaminophen might cause modifications of PDH that could induce autoantibody [AMA] formation and that drugs or environmental toxins may play a pathogenetic role in primary biliary cirrhosis). 22920894
Rumack B, Heard K, Green J, Albert D, Bucher-Bartelson B, Bodmer M, Sivilotti ML, Dart RC. Effect of therapeutic doses of acetaminophen (up to 4 g/day) on serum alanine aminotransferase levels in subjects consuming ethanol: systematic review and meta-analysis of randomized controlled trials. Pharmacotherapy 2012; 32: 784-91. (Systematic review of 6 controlled trials of acetaminophen in persons who drink alcohol indicated that serum ALT levels did not change between baseline and day 4 of acetaminophen therapy [4 g daily]). 22851428
Waring WS. Paracetamol (acetaminophen) overdose and acetylcysteine administration: should the United Kingdom adopt a single '150-line'? Br J Clin Pharmacol 2012; 74: 1066-7. (Letter discussing use of a single timed plasma concentration of acetaminophen [150 mg/L: ~1 mmol/L] to recommend acetylcysteine therapy after suspected acetaminophen overdose). 22835053
Kjartansdottir I, Bergmann OM, Arnadottir RS, Björnsson ES. Paracetamol intoxications: a retrospective population-based study in Iceland. Scand J Gastroenterol 2012; 47: 1344-52. (Analysis of diagnostic reegistry of the National University Hospital of Iceland between 2004-2009 found a decline in rate of acetaminophen overdoses and only 7 cases of severe hepatotoxicity [1 death], liver injury being more common with accidental overdose, older age and alcohol use). 22827594
Suk KT, Kim DJ, Kim CH, Park SH, Yoon JH, Kim YS, Baik GH, et al. A prospective nationwide study of drug-induced liver injury in Korea. Am J Gastroenterol 2012; 107: 1380-7. (Among 371 cases of drug induced liver injury seen at 17 University hospitals in Korea between 2005-2007, only 9 [2%] were attributed to acetaminophen, 6 of which were attributed to overdose). 22733303
Waring WS. Criteria for acetylcysteine treatment and clinical outcomes after paracetamol poisoning. Expert Rev Clin Pharmacol 2012; 5: 311-8. (Different cut-offs on the lines on the Prescott normogram are used as criteria to administer acetylcysteine after acetaminophen overdose; among 1191 patients with overdose, 16% had levels above 200, 24% above 150 and 39% above 100 mg/L; but acute liver injury occurred in 3.7% vs 2.3% vs 1.9% of patients). 22697593
Ogilvie JD, Rieder MJ, Lim R. Acetaminophen overdose in children. CMAJ 2012; 184: 1492-6. (22 day old boy was given the incorrect dose of liquid acetaminophen [800 instead of 40 mg] in preparation of circumcision and had a blood levels of 1243 umol/L, was treated with acetylcysteine, and did well without ALT elevation or symptoms of toxicity). 22664763
Wolf MS, King J, Jacobson K, Di Francesco L, Bailey SC, Mullen R, McCarthy D, Serper M, Davis TC, Parker RM. Risk of unintentional overdose with non-prescription acetaminophen products. J Gen Intern Med 2012; 27: 1587-93. (Structured interviews with 500 patients in US internal medicine practices found that 24% would use acetaminophen in doses above 4 g daily depending in part of the over-the-counter product being considered). 22638604
McQuade DJ, Dargan PI, Keep J, Wood DM. Paracetamol toxicity: What would be the implications of a change in UK treatment guidelines? Eur J Clin Pharmacol 2012; 68: 1541-7. (Cost effective analysis suggesting that use of a single timed plasma acetaminophen concentration [150 mg/L] rather than two levels [100 or 200 mg/L] and clinical assessment of risk was optimal in guiding use of acetylcysteine for acetaminophen overdose). 22527349
Craig DG, Zafar S, Reid TW, Martin KG, Davidson JS, Hayes PC, Simpson KJ. The sequential organ failure assessment (SOFA) score is an effective triage marker following staggered paracetamol (acetaminophen) overdose. Aliment Pharmacol Ther 2012; 35: 1408-15. (Based upon analyses of 138 patients with acetaminophen overdose, SOFA was superior to MELD in predicting spontaneous survival at 72 and 96 hours after overdose). 22524320
Argentieri J, Morrone K, Pollack Y. Acetaminophen and Ibuprofen overdosage. Pediatr Rev 2012; 33: 188-9. (Short review of metabolism, indications, and appropriate dosages of acetaminophen and ibuprofen in children and the clinical features and management of overdose of each). 22474118
Martinez RM, Nordt SP, Cantrell FL. Prescription acetaminophen ingestions associated with hepatic injury and death. J Community Health 2012; 37: 1249-52. (Analysis of California Poison Control database [2001-2010] for cases of prescription acetaminophen overdose with hepatic injury identified 40 cases [2 deaths, 1 liver transplant], most commonly with combinations of 500 mg of acetaminophen with hydrocodone or oxycodone and often with addition of an over-the-counter acetaminophen product). 22466137
Heard K, Bui A, Mlynarchek SL, Green JL, Bond GR, Clark RF, Kozer E, et al. Toxicity From Repeated Doses of Acetaminophen in Children: Assessment of Causality and Dose in Reported Cases. Am J Ther 2014 21: 174-83. (Systematic review of literature of cases of acetaminophen hepatotoxicity in children associated with repeated dosing indicated that injury was associated only dosing over above the recommended daily dose [<75 mg/kg]). 22407198
Thornton SL, Minns AB. Unintentional chronic acetaminophen poisoning during pregnancy resulting in liver transplantation. J Med Toxicol 2012; 8: 176-8. (22 year old woman in 2nd trimester of pregnancy took acetaminophen in doses of ~6 g daily for 2 weeks and presented with acute liver failure [initial bilirubin 2.8 mg/dL, ALT 1436 U/L, INR 1.6], progressive to stage 4 encephalopathy and undergoing successful liver transplantation; however fetus developed progressive enlargement of brain ventricles and was lost at 17 days after transplant). 22415886
Heard K, Green J. Acetylcysteine therapy for acetaminophen poisoning. Curr Pharm Biotechnol 2012; 13: 1917-23. (Review and history of major controversies surrounding development, use and recommendations on acetylcysteine therapy of acetaminophen overdose). 22352734
Voigt MD. Predicting death in patients with acetaminophen-induced acute liver failure: the King's College Hospital model is on the SOFA, not the mat. Liver Transpl 2012; 18: 384-6. (Editorial on use of SOFA, King's College criteria or MELD for predicting death from acetaminophen induced acute liver failure). 22253086
Bond GR, Ho M, Woodward RW. Trends in hepatic injury associated with unintentional overdose of paracetamol (Acetaminophen) in products with and without opioid: an analysis using the National Poison Data System of the American Association of Poison Control Centers, 2000-7. Drug Saf 2012; 35: 149-57. (Analysis of the US National Poison Data System [2000-2007] identified ~120,000 cases of overdose with acetaminophen-opioid combination, reports increasing 70% over the time period and 1614 [1.3%] having mild liver injury [ALT >100 U/L] and 1115 [1%] severe [ALT >1000 U/L], with 165 deaths and 9 liver transplants; at the same time, ~127,000 cases were identified with acetaminophen alone, reports increasing by 44% and mild liver injury occurring in 2091 [1.6%] and severe in 2583 [2%] with 267 deaths and 23 liver transplants; thus, poisonings have increased faster than overall use, particularly those associated with combination prescription products). 22149359
Hawton K, Bergen H, Simkin S, Dodd S, Pocock P, Bernal W, Gunnell D, et al. Long term effect of reduced pack sizes of paracetamol on poisoning deaths and liver transplant activity in England and Wales: interrupted time series analyses. BMJ 2013; 346: f403. (In 1998, legislation in the UK placed resistrictions on pack sizes of acetaminophen which was followed by a fall in deaths due to acetaminophen overdose [both suicidal and unintentional] by 43% and reduction in listings for transplant by 61%, but a minimal [not significant] decline in actual transplants for acetaminophen overdose).
Antoine DJ, Dear JW, Lewis PS, Platt V, Coyle J, Masson M, Thanacoody RH, et al. Mechanistic biomarkers provide early and sensitive detection of acetaminophen-induced acute liver injury at first presentation to hospital. Hepatology 2013; 58: 777-87. (Testing plasma from 129 patients presenting after an acute acetamenophen overdose [with levels that warranted acetylcysteine therapy] showed elevations in miR-122, HMGB1 and K18 well before rises in ALT, which were predictive of subsequent liver injury and thus early, prognostic markers). 23390034
Gulmez SE, Larrey D, Pageaux GP, Lignot S, Lassalle R, Jové J, Gatta A, et al. Transplantation for acute liver failure in patients exposed to NSAIDs or paracetamol (acetaminophen): the multinational case-population SALT study. Drug Saf 2013; 36: 135-44. (Case population study of adults listed for transplantation between 2005 and 2007 at 52 transplant centers in Europe; among 9479 patients, 600 were registered for acute liver failure, 192 of whom had been exposed to acetaminophen [111: 18.5% with overdose]). 23325533
James LP, Chiew A, Abdel-Rahman SM, Letzig L, Graudins A, Day P, Roberts D. Acetaminophen protein adduct formation following low-dose acetaminophen exposure: comparison of immediate-release vs extended-release formulations. Eur J Clin Pharmacol 2013; 69: 851-7. (Acetaminophen protein adducts were detected in serum within hours of ingestion of low dose acetaminophen [either immediate- or extended-release], but at levels [<0.1 nmol/mL] far below those associated with acetaminophen induced acute liver failure [>1 nmol/mL]). 23052410
Possamai LA, McPhail MJ, Quaglia A, Zingarelli V, Abeles RD, Tidswell R, Puthucheary Z, et al. Character and temporal evolution of apoptosis in acetaminophen-induced acute liver failure. Crit Care Med 2013; 41: 2543-50. (Patients with acute liver failure had high initial levels of total and caspase-cleaved cytokeratin-18 [biomarkers for apoptosis], which fell rapidly with recovery). 23949472
McGill MR, Jaeschke H. Apoptosis or necrosis in acetaminophen-induced acute liver failure? New insights from mechanistic biomarkers*. Crit Care Med 2013; 41: 2653-4. (Editorial in response to Possamai [2013]). 24162681
Hewett DG, Shields J, Waring WS. Missed paracetamol (acetaminophen) overdose due to confusion regarding drug names. Curr Drug Saf 2013; 8: 203-6. (Patient with an intentional overdose of acetaminophen referred to it as "Advil" for which reason acetylcysteine therapy was delayed). 23914754
De-Giorgio F, Lodise M, Chiarotti M, d'Aloja E, Carbone A, Valerio L. Possible Fatal Acetaminophen intoxication with atypical clinical presentation. J Forensic Sci 2013: 58: 1397-400. (63 year old woman developed hemorrhagic bullae, rhabdomyolysis, disseminated intravascular coagulation and acute renal failure [direct bilirubin 2.3 mg/dL, ALT 67 U/L, CPK 4462 U/K, creatinine 5.3 mg/dL], toxicology screening demonstrating elevated acetaminophen levels [78 mg/L] and autopsy showing steatosis, hepatitis and focal necrosis). 23822653
Rangnekar AS, Ellerbe C, Durkalski V, McGuire B, Lee WM, Fontana RJ. Quality of life is significantly impaired in long-term survivors of acute liver failure and particularly in acetaminophen-overdose patients. Liver Transpl 2013; 19: 991-1000. (Among 282 adults who survived acute liver failure spontaneously [157] or with liver transplantation [125], quality of life assessments 1-2 years later showed lower general health scores than population controls, with lowest values among spontaneous survivors of acetaminophen overdose). 23780824
Franko KR, Mekeel KL, Woelkers D, Khanna A, Hemming AW. Accidental acetaminophen overdose results in liver transplant during second trimester of pregnancy: a case report. Transplant Proc 2013; 45: 2063-5. (22 year old woman took high doses of APAP for dental pain during her 2nd trimester of pregancy and presented with acute liver failure and underwent emergency liver transplantation; 17 days later the fetus was lost; same case as Thornton [2012]). 23769109
Zhou L, Maviglia SM, Rocha RA. The ability of a retrospective review ofelectronic health records to fully capture the frequency of supratherapeuticdosing of acetaminophen--reply. JAMA Intern Med 2013; 173: 1036. (Estimated rates of regular use of aspirin [19%] and NSAIDS [12%] in the general, US adult population in 2010 from the National Health Interview Survey, representing a 57% [aspirin] and 41% [NSIADs] increase since 2005; use was higher in whites and with increasing age). 23752971
Leonis MA, Alonso EM, Im K, Belle SH, Squires RH; Pediatric Acute Liver Failure Study Group. Chronic acetaminophen exposure in pediatric acute liver failure. Pediatrics 2013; 131: e740-6. (Among 666 children with acute liver failure in a prospective database, 85 [13%] had a single dose exposure to acetaminophen and 83 [13%] chronic exposure; the two groups had similar clinical features [ALT 5140 vs 2384 U/L], but chronic exposure cases were younger [mean age 3.5 vs 15 years], less likely female [46% vs 82%], and more likely to die [12% vs 2%], however only 22% of them were diagnosed as acetaminophen overdose [37% were "indeterminant"]). 23439908
Green JL, Heard KJ, Reynolds KM, Albert D. Oral and intravenous acetylcysteine for treatment of acetaminophen toxicity: a systematic review and meta-analysis. West J Emerg Med 2013; 14: 218-26. (Metaanlysis of published literature on oral vs iv acetylcysteine for treatment and prevention of acetaminophen toxicity found similar rates of subsequent hepatitis [12.6% vs 13.2%], failures correlating best with delay in therapy, but no direct comparisons). 23687539
Court MH, Freytsis M, Wang X, Peter I, Guillemette C, Hazarika S, Duan SX, et al; Acute Liver Failure Study Group. The UDP-glucuronosyltransferase (UGT) 1A polymorphism c.2042C>G (rs8330) is associated with increased human liver acetaminophen glucuronidation, increased UGT1A exon 5a/5b splice variant mRNA ratio, and decreased risk of unintentional acetaminophen-induced acute liver failure. J Pharmacol Exp Ther 2013; 345: 297-307. (Among 260 patients with acute liver failure tested for UDP-glucuronosyltransferase [UGT] 1A polymorphism rs8330, a higher frequency of the c.2042C>G variant [enhanced glucuronidation] was found among those with unintentional [29%] than those with intentional acetaminophen overdose [46%] or other causes [42%] or matched population controls). 23408116
Kuehn BM. FDA: Acetaminophen may trigger serious skin problems. JAMA 2013; 310: 785. (Discussion of FDA warning that acetaminophen may cause Stevens Johnson Syndrome [SJS] or toxic epidermal necrolysis [TEM], a review identifying at least 91 cases, some with no other exposures and others with a positive rechallenge). 23982356
Manchanda A, Cameron C, Robinson G. Beware of paracetamol use in alcohol abusers: a potential cause of acute liver injury. N Z Med J 2013; 126: 80-4. (Commentary suggesting that the syndrome of acute serious liver injury from chronic therapeutic use of acetaminophen in alcoholic patients is underrecognized and not adequately assessed in prospective studies). 24157994
Bunchorntavakul C, Reddy KR. Acetaminophen-related hepatotoxicity. Clin Liver Dis. 2013; 17: 587-607, viii. (Comprehensive review of liver injury caused by acetamenophen with discussion of pathogenesis, epidemiology, risk factors, clinical manifestations, diagnosis, management and role of liver transplantation). 24099020
Lee WM. Drug-induced acute liver failure. Clin Liver Dis 2013; 17: 575-86, viii. (Overview of acute liver failure caused by medications which accounts for more than half of cases in recent prospective US registries; among 2000 cases in an adult registry, 916 [46%] were due to acetaminophen and 220 [10%] to other medications; N-acetylcysteine may be beneficial for both forms of acute injury). 24099019
James LP, Gill P, Simpson P. Predicting risk in patients with acetaminophen overdose. Expert Rev Gastroenterol Hepatol 2013; 7: 509-12. (Commentary on use of biomarkers to predict acetaminophen hepatotoxicity and recent study by Anoine [2013], stressing the need for a very high negative predictive value for any test result to guide management [withholding acetylcysteine therapy]). 23984999
Duffull SB, Isbister GK. Predicting the requirement for N-acetylcysteine in paracetamol poisoning from reported dose. Clin Toxicol (Phila) 2013; 51: 772-6. (Among 1571 hospital admissions [1303 different patients] for acetaminophen overdose with a patient reported dose and known time of ingestion, acetaminophen levels were above the normogram line [150/1000] in 337 and 300 received acetylcysteine found the reported dose a strong predictor, particularly if above 50 g). 23964853
Sanaei-Zadeh H. Reliability of the reported ingested dose for predicting the requirement of N-acetylcysteine in paracetamol overdose patients. Clin Toxicol (Phila) 2013; 51: 1239. (Letter in response to Dufful [2013] pointing out other publications on the issue of reliability of patient reported dose of acetaminophen). 24138504
Thulin P, Nordahl G, Gry M, Yimer G, Aklillu E, Makonnen E, Aderaye G, et al. Keratin-18 and microRNA-122 complement alanine aminotransferase as novel safety biomarkers for drug-induced liver injury in two human cohorts. Liver Int 2013 Sep 11. [Epub ahead of print] (Analysis of serum samples from patients given maximum recommended dose of acetaminophen [Watkins 2006] found elevations in cytokeratin-18 markers [M65] and miR-122 arising before increases in ALT in serum and reaching higher relative values). 24118944
Civan JM, Navarro V, Herrine SK, Riggio JM, Adams P, Rossi S. Patterns of acetaminophen use exceeding 4 grams daily in a hospitalized population at a tertiary care center. Gastroenterol Hepatol (N Y) 2014; 10: 27-34. (Analysis of inpatient electronic medical records from a single tertiary care hospital from 2008 to 2010 for acetaminophen doses identified 43,761 patients given acetaminophen, only 2.6% of whom received more than 4 g per day, often caused by use of multiple acetaminophen containing products). 24799836
McGill MR, Cao M, Svetlov A, Sharpe MR, Williams CD, Curry SC, Farhood A, et al. Argininosuccinate synthetase as a plasma biomarker of liver injury after acetaminophen overdose in rodents and humans. Biomarkers 2014; 19: 222-30. (Argininosuccinate synthetase was found to increase early in the course of liver injury due to acetaminophen in rodents; testing of patients with liver injury from acetaminophen found high levels of ASS mirroring increases in ALT). 24597531
Mendizabal M, Marciano S, Videla MG, Anders M, Zerega A, Balderramo DC, Chan D, et al. Changing etiologies and outcomes of acute liver failure: perspectives from 6 transplant centers in Argentina. Liver Transpl 2014; 20: 483-9. (Retrospective analysis of cases of acute liver failure admitted to 6 liver transplant centers in Argentina between 2005 and 2011 identified 154 cases, 16 [10%] were attributed to drugs or toxins, but none to acetaminophen overdose). 24425668
Court MH, Peter I, Hazarika S, Vasiadi M, Greenblatt DJ, Lee WM; Acute Liver Failure Study Group. Candidate gene polymorphisms in patients with acetaminophen-induced acute liver failure. Drug Metab Dispos 2014; 42: 28-32. (Analysis of several candidate gene polymorphisms in patients with acute liver failure from intentional [n=78] or unintentional [n=79] acetaminophen overdose or other causes [n=103] found no statistically significant associations, although polymorphisms of CPY 3A5 and CD44 were somewhat overexpressed in acetaminophen cases). 24104197
Karczmarek-Borowska B, Drzymała M, Golon K. [Hepatotoxicity of acetaminophen in a patient treated with capecitabine due to breast cancer]. Pol Merkur Lekarsk 2014; 36: 348-51. Polish. (Patient being treated with capecitabine for breast cancer developed liver dysfunction after taking acetaminophen [5.5 g daily for 3 days] for a viral infection). 24964515
Kang MH, Villablanca JG, Glade Bender JL, Matthay KK, Groshen S, Sposto R, Czarnecki S, et al. Probable fatal drug interaction between intravenous fenretinide, ceftriaxone, and acetaminophen: a case report from a New Approaches to Neuroblastoma (NANT) Phase I study. BMC Res Notes 2014: 7: 256. (7 year old boy with refractory neuroblastoma received experimental therapy with fenretinide and developed fever [day 4] followed by acute liver failure [peak bilirubin 22.8 mg/dL, ALT 1588 U/L, LDH 4231 U/L] with coagulopathy, ascites and lactic acidosis autopsy showing coagulative necrosis, attributed to interaction of acetaminophen, ceftriaxone and fenretinide). 24755475
Heard K, Rumack BH, Green JL, Bucher-Bartelson B, Heard S, Bronstein AC, Dart RC. A single-arm clinical trial of a 48-hour intravenous N-acetylcysteine protocol for treatment of acetaminophen poisoning. Clin Toxicol (Phila) 2014; 52: 512-8. (Among 309 patients with acetaminophen overdose presenting within 24 hours with potentially toxic serum levels who were treated with a 48 hour regimen of intravenous NAC, 18% developed ALT levels above 1000 U/L and one died). 24708414
Bucaretchi F, Fernandes CB, Branco MM, De Capitani EM, Hyslop S, Caldas JP, Moreno CA, Porta G. Acute liver failure in a term neonate after repeated paracetamol administration. Rev Paul Pediatr 2014; 32: 144-8. (26 year old male neonate was given acetaminophen orally for 3 days [10 mg/kg every 4 hours] by his breastfeeding mother who was also taking acetaminophen and presented with shock, jaundice and hepatomegaly [bilirubin 9.6 mg/dL, ALT 1087, INR 7.9, pH 7.21, glucose 18 mg/dL, ammonia 308 µg/dL], recovering with supportive measures and NAC with normal subsequent laboratory tests and neuropsychomotor development). 24676202
Michaut A, Moreau C, Robin MA, Fromenty B. Acetaminophen-induced liver injury in obesity and nonalcoholic fatty liver disease. Liver Int 2014; 34: e171-9. (Review of acetaminophen induced liver injury in obesity or nonalcoholic fatty liver disease mentions that results in animal models have been contradictory and there is no known association of increased susceptibility to liver injury from acetaminophen and body weight or fatty liver despite theoretical reasons why this might be so). 24575957
dela Cruz Ubaldo C, Hall NS, Le B. Postmarketing review of intravenous acetaminophen dosing based on Food and Drug Administration prescribing guidelines. Pharmacotherapy 2014; 34 Suppl 1: 34S-39S. (Retrospective analysis of 300 hospitalized patients who received intravenous acetaminophen for pain, found inappropriate dosing in 59 patients [20%], mostly due to not reducing dose for weight less than 50 Kg or continuing therapy for more than 24 hours; no serious adverse events were identified however). 25521845
Bateman DN, Dear JW, Carroll R, Pettie J, Yamamoto T, Elamin ME, Peart L, et al. Impact of reducing the threshold for acetylcysteine treatment in acute paracetamol poisoning: the recent United Kingdom experience. Clin Toxicol (Phila) 2014; 52: 868-72. (UK recommendations for acetaminophen levels qualifying for NAC therapy of overdose patients changed in 2012 from 150 [the US recommended levels] to 100 mg/dL and resulted in a marked increase in hospitalizations, use of NAC and medical costs with little evidence of improved outcomes). 25200454
Quartuccio L, Maset M, Soardo G, Avellini C, De Vita S. Acetaminophen-induced liver injury in a woman with febrile flare of systemic lupus erythematosus. J Clin Rheumatol 2014; 20: 349-51. (44 year old woman with systemic lupus developed rash and liver injury after being treated for fever with ciprofloxacin, amoxicillin/clavulanate and acetaminophen [4 g daily for 5 days] [bilirubin normal, ALT peak 1425 U/L, GGT 830 U/L, Alk P not given, INR normal], a liver biopsy suggesting acetaminophen injury and recovery with NAC and high dose prednisone). 25160028
Ward J, Kanchagar C, Veksler-Lublinsky I, Lee RC, McGill MR, Jaeschke H, Curry SC, Ambros VR. Circulating microRNA profiles in human patients with acetaminophen hepatotoxicity or ischemic hepatitis. Proc Natl Acad Sci U S A 2014; 111: 12169-74. (Testing serum and urine from 47 patients with acetaminophen overdose showed a positive correlation with number of microRNAs elevated in serum and ALT levels, usually rising before ALT elevations and demonstrating different patterns compared with ischemic liver injury). 25092309
Heard K, Green JL, Anderson V, Bucher-Bartelson B, Dart RC. A randomized, placebo-controlled trial to determine the course of aminotransferase elevation during prolonged acetaminophen administration. BMC Pharmacol Toxicol 2014; 15: 39. (Among 252 healthy outpatient volunteers treated with acetaminophen [4 g daily] or placebo for 16 days, ALT elevations occurred in 48 [23%] on acetaminophen vs 1[2%] on placebo and were above normal in 18 [9%] vs 1 [2%] and above twice normal in 6 [3%] vs none, with peak values at days 7-10 [highest 191 U/L]; continuation of acetaminophen to 40 days was followed by fall of values into the normal range in all except one patient). 25047090
Hedeland RL, Andersen J, Askbo N, Iskandar A, Jørgensen MH. Early predictors of severe acetaminophen-induced hepatotoxicity in a paediatric population referred to a tertiary paediatric department. Acta Paediatr 2014; 103: 1179-86. (Among 25 Danish children [22 girls, ages 11-16 years] with suicidal acetaminophen overdose and hepatotoxicity, acetaminophen intake ranged from 6.5 to 50 g and did not correlate with severity of injury; all recovered and only one had transient encephalopathy). 25041517
Curtis RM, Sivilotti ML. A descriptive analysis of aspartate and alanine aminotransferase rise and fall following acetaminophen overdose. Clin Toxicol (Phila) 2015; 53: 849-55. (Among 68 adults with acetaminophen overdose and hepatotoxicity, ALT and AST values rose and peaked together, but AST fell more rapidly than ALT [half-life of 15 vs 40 hours]). 26294195
Suzuki A, Yuen NA, Ilic K, Miller RT, Reese MJ, Brown HR, Ambroso JI, et al. Comedications alter drug-induced liver injury reporting frequency: Data mining in the WHO VigiBase™. Regul Toxicol Pharmacol 2015; 72: 481-90. (Analysis of a large database of cases of acetaminophen, isoniazid, valproate and amoxicillin/clavulanic acid induced liver injury found variation in frequency by specific comedications being taken). 25988394
Beger RD, Bhattacharyya S, Yang X, Gill PS, Schnackenberg LK, Sun J, James LP. Translational biomarkers of acetaminophen-induced acute liver injury. Arch Toxicol 2015; 89: 1497-522. (Review of results of studies of proteomics, transcriptomics and metabolomics to discover biomarkers to aid in diagnosis and management of acute acetaminophen hepatotoxicity focusing upon protein adducts for accurate diagnosis and microRNAs for prognosis and monitoring response to NAC and recovery). 25983262
Mengual-Moreno E, Lizarzábal-García M, Ruiz-Soler M, Silva-Suarez N, Andrade-Bellido R, Lucena-González M, Bessone F, et al. [Case reports of drug-induced liver injury in a reference hospital of Zulia state, Venezuela]. Invest Clin 2015; 56: 3-12. Spanish. (Among 13 patients presenting with drug induced liver injury at a Venezuelan hospital over a one year period, 2 were attributed to acetaminophen, both presenting a month after starting with mild-to-moderate serum aminotransferase elevations only, both resolving upon stopping). 25920181
Frey SM, Wiegand TJ, Green JL, Heard KJ, Wilkins DG, Gorodetsky RM, Dart RC. Confirming the causative role of acetaminophen in indeterminate acute liver failure using acetaminophen-cysteine adducts. J Med Toxicol 2015; 11: 218-22. (26 year old woman with recurrent severe acute hepatitis denied significant acetaminophen ingestion, but had typical clinical course and acetaminophen-cysteine adducts were detected in serum taken 4 days after presentation, securing the diagnosis and leading to her admitting to purposeful intake). 25896948
Alonso EM, James LP, Zhang S, Squires RH; Pediatric Acute Liver Failure Study Group. Acetaminophen Adducts Detected in Serum of Pediatric Patients With Acute Liver Failure. J Pediatr Gastroenterol Nutr 2015; 61: 102-7. (Among 393 children with acute liver failure, acetaminophen-cysteine adducts were detected in 50 of 58 [86%] with suspected acetaminophen overdose, 21 of 190 [11%] with indeterminant cause and 8 of 145 [5.5%] with specific causes). 25859823
Harimoto N, Wang H, Ikegami T, Takeishi K, Itoh S, Yamashita YI, Yoshizumi T, et al. Education and imaging. Hepatology: Rare Stevens-Johnson syndrome and vanishing bile duct syndrome induced by acetaminophen, requiring liver transplantation. J Gastroenterol Hepatol 2015; 30: 656. (40 year old woman developed Stevens Johnson syndrome attributed to acetaminophen [no information given on dose or timing or other exposures: biliribin 27.9 mg/dL, ALT 17 U/L, Alk P 894 U/L, INR 1.3], undergoing living donor liver transplantation, explant showing vanishing bile duct syndrome). 25776963
Ioannides SJ, Siebers R, Perrin K, Weatherall M, Crane J, Travers J, Shirtcliffe P, Beasley R. The effect of 1g of acetaminophen twice daily for 12 weeks on alanine transaminase levels--A randomized placebo-controlled trial. Clin Biochem 2015; 48: 713-5. (Among 94 adults with asthma treated wiith acetaminophen [2 g daily] or placebo for 12 weeks, ALT elevations above 3 times ULN arose in 1 subject in both groups, and mean ALT levels were minimally increased with acetaminophen [from 23.6 to 25.4 U/L], but not placebo [from 19.5 to 19.0 U/L]). 25899926
Hayward KL, Powell EE, Irvine KM, Martin JH. Can Paracetamol Acetaminophen) be administered to Patients with Liver Impairment? Br J Clin Pharmacol 2015 Oct 13. [Epub ahead of print] (Review of the safety of acetaminophen in patients with liver dysfunction mentions that serum levels are slightly higher in patients with cirrhosis and recommends more conservative dosing in patients with significant liver disease). 26460177
Graudins A. Paracetamol poisoning in adolescents in an Australian setting: not quite adults. Emerg Med Australas 2015; 27: 139-44. (Among 187 adolescents presenting with acetaminophen overdose at 3 Australian medical centers during a 4 year period, 89% were girls, 53% ingestied acetaminophen alone and 96% were intentional overdoses; 107 received NAC, none died on underwent liver transplantation; liver injury not mentioned). 25752743
Goldberg DS, Forde KA, Carbonari DM, Lewis JD, Leidl KB, Reddy KR, Haynes K, et al. Population-representative incidence of drug-induced acute liver failure based on an analysis of an integrated health care system. Gastroenterology 2015; 148: 1353-61. (Among more than 4 million adults participating in an integrated health care system in Northern California, 62 developed possible or definite acute liver failure [ALF] of which 32 [52%] were due to drugs, including acetaminophen [18: 56%], HDS [6: 19%] and various prescription drugs [8:25%] including isoniazid [n=1] and amoxicillin/clavulanate [n=1]; 6 patients had liver transplant and 4 died; estimated incidence of ALF was 1.6 per million and acetaminophen ALF 1 per million population). 25733099
Yang X, Salminen WF, Shi Q, Greenhaw J, Gill PS, Bhattacharyya S, Beger RD, et al. Potential of extracellular microRNAs as biomarkers of acetaminophen toxicity in children. Toxicol Appl Pharmacol 2015; 284: 180-7. (Comparison of microRNA profiling among 8 children with acetaminophen overdose and hepatotoxicity, to 10 children on therapeutic doses and 10 normal children demonstated increases in 8 different microRNAs with hepatic injury including miRNA-122 and -375). 25708609
Kocaaslan ND, Tuncer FB, Tutar E, Celebiler O. Acute liver failure and hepatic encephalopathy after cleft palate repair. Cleft Palate Craniofac J 2015; 52: 629-31. (12 month old boy underwent cleft palate repair and received rectal and oral acetaminophen of 96 mg/kg for one day and 60 mg/kg daily for 3 days and presented with bloody vomiting, severe hypoglycemia and liver failure [bilirubin 1.3 mg/dL, ALT 2467 U/L, INR 3.1], responding to supportive care). 25689020
Lee PJ, Shen M, Wang S, Spiegler P, Caraccio T, DeMuro JP, Malone B. Possible hepatotoxicity associated with intravenous acetaminophen in a 36-year-old female patient. P T 2015; 40: 123-32. (36 year old woman received 6 days of intravenous acetaminophen [~4 g daily] and developed marked liver injury [bilirubin 2.0 mg/dL, ALT 6600 U/L, AST 4833 U/L, Alk P normal, INR 3.8], ultimately recovering after stopping acetaminophen and administering NAC). 25673962
McGovern AJ, Vitkovitsky IV, Jones DL, Mullins ME. Can AST/ALT ratio indicate recovery after acute paracetamol poisoning? Clin Toxicol (Phila) 2015; 53: 164-7. (Among 37 patients with hepatotoxicity from acetaminophen overdose, the AST/ALT ratio of <0.5 was highly indicative of values after the peak of enzyme elevations in patients who recovered). 25652258
Holt EW, DeMartini S, Davern TJ. Acute liver failure due to acetaminophen poisoning in patients with prior weight loss surgery: a case series. J Clin Gastroentero. 2015; 49: 790-3. (Among 101 patients with acute liver failure presenting at a single California transplant center over a 3 year period, 9 of 54 subjects with acetaminophen overdose vs none of 47 with ALF of other causes had a history of weight loss surgery; course and outcome of acetaminophen related ALF was similar between those with bariatric surgery and those without, two-thirds of cases were unintentional overdose). 25551211
Lancaster EM, Hiatt JR, Zarrinpar A. Acetaminophen hepatotoxicity: an updated review. Arch Toxicol 2015; 89: 193-9. (Review of acetaminophen hepatotoxicity focusing upon pathophysiology [CYP 2E1 metabolism], risk factors [decrease in glutathione or upregulation of CYP 450], clinical presentation, management [NAC, and use of Rumack-Matthew normogram], liver support systems, liver transplantation and outcomes). 25537186
Park HJ, Kim SR, Leem DW, Moon IJ, Koh BS, Park KH, Park JW, et al. Clinical features of and genetic predisposition to drug-induced Stevens-Johnson syndrome and toxic epidermal necrolysis in a single Korean tertiary institution patients-investigating the relation between the HLA -B*4403 allele and lamotrigine. Eur J Clin Pharmacol 2015; 71: 35-41. (Among 30 cases of SJS/TEN seen at a single Korean medical referral center between 2010 and 2014, 8 were attributed to lamotrigine, 8 to allopurinol, and 3 to acetaminophen). 25327504
Rajanayagam J, Bishop JR, Lewindon PJ, Evans HM. Paracetamol-associated acute liver failure in Australian and New Zealand children: high rate of medication errors. Arch Dis Child 2015; 100: 77-80. (Among 54 cases of acute liver failure in children seen at two pediatric transplant centers in Australia [Brisbane] and New Zealand [Auckland] between 2001 and 2012, 14 were due to acetaminophen overdose, 12 in children <5 years of age and usually due to dosing error, range of doses 62 to 250 mg daily for 2 to 24 days; 3 underwent liver transplant, 2 died). 25228327
Mishima-Iwai M, Takahashi K, Yokode M, Kimura Y, Sawai Y, Ueda Y, Chiba T. Late-onset acetaminophen-induced allergic hepatitis with progression to chronicity. Hepatol Res 2015; 45: 814-7. (35 year old Japanese woman developed acute liver injury first noted 14 days after a 2-day course of acetaminophen, cefcapene and loxoprofen which progressed to an acute icteric hepatitis 6 weeks later [peak bilirubin 8.2 mg/dL, ALT 659 U/L, prothrombin index 35%] with ascites and encephalopathy responding to corticosteroids, but ALT elevations persisting with positive lymphocyte stimulation test to acetaminophen only). 25088083
Fontana RJ, Ellerbe C, Durkalski VE, Rangnekar A, Reddy RK, Stravitz T, McGuire B, et al.; US Acute Liver Failure Study Group. Two-year outcomes in initial survivors with acute liver failure: results from a prospective, multicentre study. Liver Int 2015; 35: 370-80. (Among 306 patients with acute liver failure due to acetaminophen overdose who survived for 21 days, 2 year mortality was 10.5%, but most occurred within 3 months and mortality correlated with age and severity of the acute episode [ALT levels, coma grade]). 25039930
Vliegenthart AD, Shaffer JM, Clarke JI, Peeters LE, Caporali A, Bateman DN, Wood DM, et al. Comprehensive microRNA profiling in acetaminophen toxicity identifies novel circulating biomarkers for human liver and kidney injury. Sci Rep 2015; 5: 15501. (Analysis of plasma samples from 27 patients with and 27 without organ injury due to acetaminophen overdose for microRNA found greatest increases with miR-122, -885 and -151aa and miR-122 was better than ALT in predicting severe toxicity at early time points). 26489516
Kulkarni S, Perez C, Pichardo C, Castillo L, Gagnon M, Beck-Sague C, Gereige R, et al. Use of Pediatric Health Information System database to study the trends in the incidence, management, etiology, and outcomes due to pediatric acute liver failure in the United States from 2008 to 2013. Pediatr Transplant 2015; 19 (8): 888-95. (Analysis of admissions to 16 US pediatric liver transplant centers from 2008 to 2013 identified 583 patients, 53% indeterminant, 19% acetaminophen, 9% autoimmune, 2.7% metabolic and 6.5% viral hepatitis; mortality rate only 5% and 73% survived with their native liver). 26388211
Serper M, Wolf MS, Parikh NA, Tillman H, Lee WM, Ganger DR. Risk Factors, Clinical presentation, and outcomes in overdose With acetaminophen alone or with combination products: results from the acute liver failure study group. J Clin Gastroenterol 2016; 50: 85-91. (Among 666 adults with acetaminophen overdose and acute liver failure seen between 1998 and 2012, 30% were taking acetaminophen alone, 14% with an antihistamine and 57% in a combination product with opioids; 62% of cases were unintentional which were most frequent with opioid combinations but course and outcomes were similar, transplantation within 7 days in 7%, death in 17%). 26166142
Seifert SA, Kovnat D, Anderson VE, Green JL, Dart RC, Heard KJ. Acute hepatotoxicity associated with therapeutic doses of intravenous acetaminophen. Clin Toxicol (Phila) 2016 Jan 14:1-4. [Epub ahead of print] (92 year old woman received 6 days of intravenous acetaminophen [1 g every 6 hours] for postoperative pain] and developed nausea, vomiting and epigastric pain [bilirubin 1.8 mg/dL, ALT 3914 U/L, AST 4698 U/L, INR 1.7, ammonia 60 µg/dL, APAP-CyS adducts 4 µM], responding to course of NAC). 26763284

## OTHER REFERENCE LINKS

1. Recent References on Acetaminophen: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Acetaminophen/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Acetaminophen: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Acetaminophen)